# Estrogens and Oral Contraceptives

## OVERVIEW

### Introduction

Estrogens and oral contraceptives are both associated with several liver related complications including intrahepatic cholestasis, sinusoidal dilatation, peliosis hepatis, hepatic adenomas, hepatocellular carcinoma, hepatic venous thrombosis and an increased risk of gallstones. These side effects are more common with higher doses of estrogens, as were used in the early high dose estrogen formulation of oral contraceptives, but they have also been described with use of more modern birth control pills and with low dose, estrogen hormonal replacement therapy.

### Background

Synthetic estrogens for regulation of menstrual cycles and hormonal replacement therapy were developed in the early 1950s and came into increasing use in thereafter. Oral contraceptives (OCCs) were approved for use in the United States in 1960 and became widely used. Initial OCCs (first generation) used somewhat high doses of estrogens (50 μg of mestranol or 20 to 50 μg of ethinyl estradiol) in combination with a progestin and had appreciable rates of estrogenic side effects. Second and third generation OCCs introduced in the 1980s and 1990s have lower doses of ethinyl estradiol (15 to 35 μg) and more modern forms of progestins (norgestrel, desogestrel and others), which have been associated with lower rates of estrogenic and other adverse side effects. Hormonal replacement therapy became increasing popular in the 1980s and 1990s. Both estrogen only and combination forms of hormonal replacement therapy were used. In women with a uterus, combination hormonal replacement therapy was recommended usually combining a conjugated equine estrogen with medroxyprogesterone. The estrogen doses used in hormonal replacement therapy were 5 to 6 times lower than the equivalent ethinylestradiol doses used in OCCs. The popularity of hormonal replacement therapy decreased in the late 1990s when prospective studies demonstrated excess morbidity and mortality associated with replacement therapy in postmenopausal women. Commercially available OCCs include monophasic, biphasic, triphasic, extended cycle and progestin only formulations. Hormonal replacement therapy usually employs conjugated equine estrogen in doses of 1.25 mg per day, with medroxyprogesterone late in the menstrual cycle.

### Hepatotoxicity

While early formulations of OCCs were associated with frequent serum enzyme elevations, current formulations and hormonal replacement therapy have not been linked to ALT or alkaline phosphatase elevations at rates any higher than occur with placebo. Estrogens and OCCs can cause mild inhibition of bilirubin excretion, leading to jaundice in patients with inherited forms of bilirubin metabolism such as the Dubin Johnson syndrome. More importantly, estrogens and OCCs can induce a clinically apparent cholestatic liver injury which typically arises during the first few cycles of therapy, and rarely after the six months (Case 1). The onset is typically insidious with fatigue and pruritus, followed by nausea, dark urine and jaundice. Serum enzyme elevations are usually mixed or cholestatic, although very early during the injury, ALT levels can be markedly elevated (5- to 20-fold). The characteristic pattern, however, is bland intrahepatic cholestasis and liver biopsy shows little inflammation or hepatocyte necrosis. Resolution may be delayed (Case 2), but estrogens have not been definitely linked to chronic injury, vanishing bile duct syndrome or acute liver failure. Women with OCC induced cholestasis often have a history of idiopathic cholestasis of pregnancy and there is likely a genetic component, most commonly with variants in the bile salt export pump (BSEP, ABC B11). Estrogens and particularly combinations of estrogens and progestins have been linked to episodes of marked serum aminotransferase elevations without symptoms, jaundice or cholestasis. The abnormalities resolve quickly with stopping the hormonal treatment. This syndrome may be more frequent with progestins than with estrogens alone.

Estrogens and OCCs have also been linked to hepatic tumors, both benign and malignant. Numerous reports of hepatic adenomas have been linked to estrogen and OCC use, typically arising after several years of use and presenting either with pain, liver mass or rupture with hemoperitoneum (Case 3). In population based surveys, the risk of developing hepatic adenomas on OCCs is estimated to be 0.5% per year. In some instances, malignant transformation and hepatocellular carcinoma have been found. Benign tumors may regress to some extent with stopping estrogens, but others require intervention. Estrogens may also promote the growth of other benign liver tumors, such as focal nodular hyperplasia, hemangiomas, and hamartomas.

Hepatocellular carcinoma has been linked to use of oral contraceptives in several case reports and case controlled studies. However, in larger studies and population based analyses, oral contraceptives have not been clearly linked to liver cancer. Hepatocellular carcinoma is extremely rare in young women without accompanying liver disease, and even if oral contraceptives increase the risk of this cancer by 2- to 3-fold, it remains extremely rare.

Use of oral contraceptives has also been linked to an increase in venous thrombosis and cases of hepatic venous thrombosis or Budd Chiari syndrome (Case 4). Women who develop this complication are often found to have other risk factors for venous thromboses such as Protein C or Protein S deficiency or Factor V Leiden. Portal vein thrombosis has also been reported with oral contraceptive use.

Chronic use of oral contraceptives is associated with sinusoidal dilatation, a finding on liver biopsy of uncertain significance. Extreme sinusoidal dilatation associated with venous lakes and propensity for hepatic rupture is referred to as peliosis hepatis, which can be associated with symptoms and hepatic rupture. Oral contraceptive use has been associated with rare instances of peliosis hepatis, but the association a striking dilation of sinusoids with venous lakes has been rarely reported with oral contraceptive use. Stopping oral contraceptives has occasionally been associated with regression in the severity of peliosis.

Both oral contraceptives and chronic hormonal replacement therapy are also associated with a slight increased rate of gallbladder disease, typically occurring during the first few years of estrogen use.

Likelihood score: A (well known cause of various forms of clinically apparent liver injury).

### Mechanism of Injury

Cholestasis due to estrogens and OCCs appears to be related to inhibition of bilirubin and bile acid secretion related to effects of estrogens on the orphan nuclear receptors that modulate bile acid and bilirubin metabolism. Women with cholestasis caused by OCCs often have a history of cholestasis of pregnancy (with jaundice and/or pruritus), and genetic variations in bile acid transporter genes (ABC B4, B11 and C2) are frequent. In addition, women who develop hepatic adenomas on OCCs are often heterozygous for gene variations associated with multiple hepatic adenomas such as in hepatic nuclear factor 1 alpha (HNF1-alpha).

### Outcome and Management

The cholestasis associated with OCCs is typically mild and resolves rapidly with stopping. Some cases, however, are protracted and associated with severe pruritus with or without marked jaundice. The efficacy of ursodiol in treating the cholestasis of pregnancy makes this approach appropriate in women who develop cholestasis due to OCCs in whom symptoms are problematic; the dosage is 12 to 15 mg/kg/day and it should be continued until symptoms and major blood test abnormalities have resolved. Corticosteroids should not be used. Recurrence of cholestasis with restarting OCCs is typical, although lower dose formulations may be found that do not trigger the response. Management of hepatic tumors related to OCCs is complex. In many instances, merely stopping oral contraceptives is followed by regression in the tumor size, but surgery may be required for larger tumors and those in which malignant transformation is believed to a risk.

See also Progesterone and the Progestins

## CASE REPORTS

### Case 1. Cholestasis due to birth control pills.(1)

A 28 year old woman developed pruritus within 4 days of starting oral contraceptives and stopped them after a week. One week later (14 days after starting), she had darkening of the urine and 4 weeks later was found to the jaundiced. She was taking no other medications and had no risk factors for viral hepatitis. Important in her past medical history were episodes of jaundice and pruritus during two pregnancies. The jaundice arose during the fifth month of her second and the sixth week of her third pregnancies with peak bilirubin values of 3.5 and 3.8 mg/dL and prominence of pruritus. The cause of jaundice during her pregnancies was not identified despite extensive evaluation including laparotomy and cholecystectomy (the gallbladder was normal without stones). Thereafter, she was well until she started birth control pills. On examination, she was jaundiced but had no fever or rash. Serum bilirubin was 4.5 mg/dL, ALT 352 U/L and alkaline phosphatase 24 King Armstrong units (~2 times upper limit of normal) (Table). A liver biopsy showed intrahepatic cholestasis with minimal inflammation. Upon stopping the contraceptive pills, serum laboratory tests improved and jaundice cleared within 2 weeks. However, she continued to have pruritus for 3 months after stopping the medication. Ultimately, all symptoms and itching resolved and laboratory tests except for alkaline phosphatase were normal 6 months later.

#### Key Points

Medication: | Enovid (once daily)
Pattern: | Mixed (R=4.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 days to symptoms, 2 weeks to jaundice
Recovery: | Jaundice resolved in 2 weeks, symptoms in 3 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (KA U/L) | Bilirubin (mg/dL) | Other
| | Enovid once daily for 7 days
6 weeks | 5 weeks | 352 | 24 | 4.2 | Direct bilirubin 2.4
7 weeks | 6 weeks | 356 | 25 | 5.5 | Liver biopsy
3 months | 11 weeks | 58 | 27 | 1.2
8 months | 30 weeks | 38 | 20 | 0.8
Normal Values | | <40 | <13 | <1.2

#### Comment

A woman with a history of idiopathic cholestasis of pregnancy developed pruritus a few days after starting birth control pills, and dark urine followed by jaundice several weeks later. The ratio of ALT to alkaline phosphatase elevations suggested that the injury was "mixed," but the liver biopsy showed bland intrahepatic cholestasis with little hepatocyte necrosis or inflammation, and the symptoms were decidedly cholestatic with a prominence of pruritus that only slowly resolved.

### Case 2. Prolonged cholestasis due to birth control pills.(2)

A 22 year old woman developed jaundice and pruritus after a single 28 day cycle of oral contraceptives (L-Ovral: orgestrel 0.3 mg and ethinyl estradiol 0.03 mg) which were started shortly after a first trimester abortion. Over the next several months, she developed worsening pruritus, anorexia, nausea, fatigue and weight loss. She had no previous history of liver disease or risk factors for viral hepatitis. Her only medications were birth control pills and rarely acetaminophen for pain. Examination showed marked jaundice and multiple excoriations. The liver was enlarged and somewhat tender to palpation. Laboratory results showed bilirubin of 7.0 mg/dL, ALT 80 U/L and Alk P 170 U/L (Table). Because of persistent jaundice, she underwent endoscopic retrograde cholangiopancreatography which was normal. A liver biopsy showed intrahepatic cholestasis with minimal inflammation and bile duct proliferation. She eventually began to improve and all laboratory values were normal or near normal 6 months later.

#### Key Points

Medication: | L-Ovral (once daily for one cycle)
Pattern: | Cholestatic (R=1.7 falling to 0.9)
Severity: | 3+ (jaundice, prolonged)
Latency: | 1 month
Recovery: | 6 months
Other medications: | Occasional acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
L-Ovral once daily for 28 days
1 month | 0 | 90 | 165 | 7.0 | Pruritus and jaundice
| 2 weeks | 80 | 250 | 11.0
2 months | 4 weeks | 105 | 290 | 15.3
| 6 weeks | 110 | 405 | 17.5 | ERCP and liver biopsy
3 months | 8 weeks | 130 | 380 | 18.2
| 10 weeks | 145 | 390 | 19.5
4 months | 12 weeks | 155 | 490 | 17.5
| 14 weeks | 190 | 556 | 13.6
5 months | 4 months | 219 | 360 | 5.8
6 months | 5 months | 60 | 200 | 1.7
7 months | 6 months | 35 | 125 | 0.5
Normal Values | | <40 | <115 | <1.2

* Values and dates estimated from Figure 1.

#### Comment

Oral contraceptive induced jaundice usually arises during the first cycle of birth control pills and is typically cholestatic with mild jaundice and pruritus, resolving in 1 to 2 months. In this instance, jaundice and pruritus were prolonged and laboratory values did not return to normal or near normal for 6 months. While oral contraceptives can cause prolonged jaundice, they have not been definitely associated with vanishing bile duct syndrome or fatal liver disease.

### Case 3. Hepatic adenoma due to birth control pills.(3)

A 28 year old woman who had been on oral contraceptives (0.25 mg d-norgestrel and 0.05 mg ethinyl estradiol: Ovral) for 7 years presented with dull, but steady right upper quadrant pain lasting for two days. She had no other significant medical problems and took no medications except occasional aspirin. She rarely drank alcohol and had no risk factors for viral hepatitis or liver disease. Physical examination revealed an obvious mass in the epigastrium and right upper quadrant that appeared to involve the liver. There was no tenderness, ascites, wasting or jaundice. Laboratory results showed an alkaline phosphatase of 1038 U/L, but normal bilirubin and ALT. The sedimentation rate was 59 mm/hr and hemoglobin 10.4 g/dL. A technetium colloid liver-spleen scan showed a large liver, but no obvious masses whereas a HIDA scan showed a large hypofunctioning mass in the liver. A liver biopsy showed hepatic adenoma with sinusoidal dilatation. A hepatic arteriogram showed a large vascular tumor occupying most of the right and central lobes. Resection was not considered technically possible. Oral contraceptives were stopped and she underwent tubal ligation. During the ensuing 12 months she remained well and repeat scans showed return of liver to normal size. Alkaline phosphatase also fell to normal.

#### Key Points

Medication: | Oral contraceptives for 7 years
Pattern: | Alkaline phosphatase elevation only
Latency: | 7 years
Recovery: | Radiological resolution over 12 months
Other medications: | Aspirin

#### Comment

Hepatic adenomas are a rare, but well defined complication of long term use of oral contraceptives. They can present in three manners: (1) with sudden acute right upper quadrant pain and rupture, (2) as an abdominal mass with or without mild degrees of pain, or (3) as an incidental finding on physical examination, during unrelated abdominal surgery or on routine radiological imaging. The association of contraceptive use and hepatic adenomas has been made both epidemiologically and clinically, the clinical evidence being supported by the rarity of this tumor before the introduction of oral contraceptives, and the spontaneous resolution or shrinkage of the tumors upon withdrawal of the pill as in this case. Serum alkaline phosphatase levels are raised in some, but certainly not all women with this tumor and liver tests are typically normal. In this instance, the high alkaline phosphatase levels were probably related to the size of the tumor and its encroachment on the normal liver and biliary system. This case also demonstrates that the tumor can be managed by stopping the oral contraceptives and careful follow up. In rare instances, hepatic adenomas have later been found to show malignant transformation. There is likely a genetic basis to the development of hepatic adenomas on oral contraceptives.

### Case 4. Budd Chiari syndrome in a woman on long term oral contraceptives.(4)

A 26 year old woman presented with a three month history of abdominal and lower leg swelling associated with a 30 pound weight gain. She was on oral contraceptives which she had taken on and off for a total of 7 years. She denied history of liver disease, abdominal trauma or previous problems with venous thrombosis. Examination showed severe ascites and peripheral edema without jaundice or peripheral manifestations of chronic liver disease. She did not drink alcohol and had no history of high risk behaviors. Laboratory testing showed a normal bilirubin [0.6 mg/dL] and ALT [10 U/L] with mild elevations in alkaline phosphatase [189 U/L]. Hepatic imaging showed enlargement of the caudate lobe and evidence of hepatic venous thrombosis. Oral contraceptives were stopped and she was treated with salt restriction, diuretics, aspirin and dipyridamole. Over the next few weeks, her ascites and fluid retention resolved. She did not have recurrence of abdominal pain or ascites during a follow up period of 22 months.

#### Key Points

Medication: | Ovulen 21 (two years, previously 5 years)

#### Comment

A woman developed hepatic vein thrombosis (Budd Chiari syndrome) with a subacute presentation of fluid retention and ascites during long term oral contraceptive use. No other predisposing factors for venous thrombosis was identified, but this syndrome most frequently occurs in persons with an underlying hypercoagulable state such as a myeloproliferative disorder or acquired abnormalities of coagulation such as the lupus anticoagulant or anticardiolipin antibodies, or inherited abnormalities such as in protein C and S or abnormalities of clotting factors V and II. Thus, Budd Chiari syndrome occurring in women on oral contraceptives may represent a paradigm of drug induced liver injury, resulting from the combination of an environmental exposure (oral contraceptives) and host, genetic predisposition.

## PRODUCT INFORMATION

DRUG CLASS

Hormones and Synthetic Substitutes:

Contraceptives, Oral; Estrogens

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ESTROGEN&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CITED REFERENCES

1 Boake WC, Schade SG, Morrissey JF, Schaffner F. (1965). Intrahepatic cholestatic jaundice of pregnancy followed by Enovid-induced cholestatic jaundice. Ann Intern Med.
2 Lieberman DA, Keefe LB, Stenzel P. (1984). Severe and prolonged oral contraceptive jaundice. J Clin Gastroenterol.
3 Steinbrecher UP, Lisbona R, Huang SN, Mishkin SI. (1981). Complete regression of hepatocellular adenoma after withdrawal of oral contraceptive use. Dig Dis Sci.
4 Lewis JH, Tice HL, Zimmerman HJ. (1983). Budd-Chiari syndrome associated with oral contraceptive steroids: review of treatment of 47 cases. Dig Dis Sci.

## ANNOTATED BIBLIOGRAPHY

References updated: 30 May 2020

Abbreviations: OCC, oral contraceptives; FNH, focal nodular hyperplasia; BRIC, benign recurrent intrahepatic cholestasis.

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 555-88. (Expert review of effects of estrogens and birth control pills on the liver).
Chitturi S, Farrell GC. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 605-20. (Review of hepatotoxicity of oral contraceptive steroids including cholestasis, vascular disorders, benign tumors and hepatocellular carcinoma).
Levin ER, Vitex WS, Hammes SR. Estrogens and progestins. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-32. (Textbook of pharmacology and therapeutics).
Perez-Mera RA, Shields CE. (1962). Jaundice associated with norethindrone acetate therapy. N Engl J Med. (35 year old woman developed jaundice and abdominal pain 2 years after starting norethindrone for dysmenorrhea with bilirubin 6.5 mg/dL, biopsy showing intrahepatic cholestasis and repeat biopsy 2 months after stopping estrogen showing resolution).
Eisalo A, Jaervinen PA, Luukkainen T. (1964). Hepatic impairment during the intake of contraceptive pills: clinical trial with postmenopausal women. Br Med J. (12 postmenopausal Finnish women were treated with progesterone or estrogen or both [Lyndiol] for 28 days; on estrogen [methoxy-ethynylestradiol], ALT elevations occurred in all patients with peak ALT 260-1900 U/L, bilirubin rise to 2.4 mg/dL in 1 and Alk P rise in 1, ALT usually peaking at 21-28 days, normalizing rapidly on stopping; no change on progesterone).
Adlercreutz H, Ikonen E. (1964). Oral contraceptives and liver damage. Br Med J. (Letter in response to Eisalo et al.; mentions their own publications in Scandinavian literature, 3 cases of jaundice on OCCs, one had jaundice of pregnancy and repeated bouts of jaundice on various formulations of OCCs, degree of tolerance relating to estrogen content).
Palva IP, Mustala OO. (1964). Oral contraceptives and liver damage. Br Med J. (Five postmenopausal women were treated with OCCs [Anovlar: 4 mg norethisterone and 0.05 ethinyloestradiol]; AST levels rose in all five after 1 week with peak values 61-340 U/L, BSP raised in all and bilirubin in 2 patients; no mention of symptoms; laboratory abnormalities resolved slowly upon stopping).
Swaab LI. (1964). Oral contraceptives and liver damage. Br Med J. (Analysis in 500 women taking two forms of OCCs; among 60 women who were monitored prospectively no elevations in AST or bilirubin levels were found).
Fawcett JW, Pederson DL. (1964). Oral contraceptives and liver damage. Br Med J. (35 year old woman developed fever, rash and liver test abnormalities [bilirubin 5.9 mg/dL, ALT 260 U/L, Alk P 3 times ULN] during the 4th month of OCC use, resolving within 2 weeks, but no mention of whether OCCs were stopped).
Linthorst G. (1964). Liver function after long-term progestational treatment with and without estrogen. Br Med J. (Among 300 women treated with Lyndiol OCCs, none developed jaundice; prospective study in 50 patients treated for 14 to 43 months found no confirmed abnormalities of liver tests).
Rice-Wray E. (1964). Oral contraceptives and liver damage. Brit Med J. (In studies of 56 women receiving Lyndiol as birth control, none developed ALT abnormalities during 3 to 12 cycles of therapy).
Sotaniemi E, Kreus KE, Scheinin TM. (1964). Oral contraceptives and liver damage. Br Med J. (24 year old woman developed itching after 10 days on OCCs with subsequent jaundice [bilirubin 8.2 rising to 14.6 mg/dL, Alk P 1.5 rising to 3 times ULN, AST 40 U/L], biopsy showing intrahepatic cholestasis, resolving within 7 weeks of stopping).
Wetterberg L. (1964). Oral contraceptives and acute intermittent porphyria. Lancet. (26 year old woman with frequent attacks of porphyria developed nausea and abdominal pain on OCCs [bilirubin 0.3 mg/dL, ALT 450 U/L, normal Alk P], improved on stopping OCCs).
Borglin NE. (1965). Oral contraceptives and liver damage. Br Med J. (36 Swedish women [ages 22-44 years] with endometriosis were treated with lynoestrenol or Lyndiol for 3 months; ALT rose in 4 of 10 patients receiving Lyndiol with peak values of 42, 72, 310 and 430 U/L, resolving rapidly with stopping).
Gate JM. (1965). Oral contraceptives and liver injury. Br Med J. (Letter commenting that liver injury due to oral contraceptives may be underreported because of small studies of short term use).
Morton WA, Johnstone FR. (1965). Oral contraceptives and liver injury. Br Med J. (Editorial on the safety of OCCs; despite widespread use, the numbers of cases of frank liver injury attributed to them are few).
Boake WC, Schade SG, Morrissey JF, Schaffner F. (1965). Intrahepatic cholestatic jaundice of pregnancy followed by Enovid-induced cholestatic jaundice. Ann Intern Med. (28 year old woman developed pruritus within 4 days of starting OCCs and later jaundice despite stopping [bilirubin 5.5 mg/dL, ALT 356 U/L, Alk P 2 times ULN], resolving slowly after stopping; had history of two episodes of jaundice during pregnancies: Case 1).
Eisenstadt HB. (1965). Abnormal liver function and synthetic estrogens. JAMA. (25 year old woman developed fatigue and nausea 9 months after starting OCCs [Ortho-Novum] with normal liver tests except BSP [18%] and liver biopsy showing excess lipofuscin, symptoms resolved with stopping pill).
Cullberg G, Lundstrom R, Stenram U. (1965). Jaundice during treatment with an oral contraceptive, Lyndiol. Br Med J. (39 year old woman developed nausea and pruritus within 10 days of starting OCC [bilirubin 8.4 mg/dL, ALT 230 U/L, Alk P 8 times ULN], resolution not mentioned).
Stoll BA, Andrews JT, Motteram R, Upfill J. (1965). Oral Contraceptives and liver damage. Br Med J. (Among 4 women given OCCs [6 pills daily] for breast cancer, all developed AST elevations >200 U/L after 2 weeks of therapy and two were jaundiced; biopsies showed centrilobular cholestasis and necrosis; resolving with stopping).
Carlström H, Höglund S, Reizenstein P. (1965). Oral contraceptives and liver damage. Br Med J. (38 year old woman with history of pruritus of pregnancy developed pruritus and jaundice after starting OCCs [bilirubin 6.1 mg/dL, Alk P 2 times ULN, eosinophils 18%], resolving with stopping drug).
Larsson-Cohn U, Stenram U. (1965). Jaundice during treatment with oral contraceptive agents. Report of two cases. JAMA. (Two women, ages 44 and 28 developed pruritus within 1-2 weeks of starting OCCs [bilirubin 3.0-7.0 mg/dL, ALT 480-730 U/L and Alk P 1-2 times ULN], resolving within 2-3 weeks of stopping; one had history of cholestasis of pregnancy).
Oigaard A. (1965). Ugeskr Laeger. (21 year old woman developed jaundice within few weeks of starting OCCs [AST 107 U/L, Alk P 3 times ULN], biopsy showing intrahepatic cholestasis, slow recovery on corticosteroids).
Elliott AJ, Hendry J. (1965). Cholestatic jaundice complicating pregnancy. Recurrence after norethynodrel with ethynylestradiol (Enovid). Can Med Assoc J. (26 year old woman had marked pruritus during 3 pregnancies beginning ~6th month with jaundice that rapidly resolved with delivery; developed itching and jaundice within 2 weeks of starting OCCs [bilirubin 6.3 mg/dL, AST 50 U/L, Alk P 13.7 KA], resolving rapidly on stopping).
Baines GF. (1965). Jaundice in a patient taking norethisterone compound tablets. Lancet. (Woman developed jaundice during second cycle of OCCs [bilirubin 7.5 mg/dL], resolving rapidly on stopping).
Becker FT. (1965). Porphyria cutanea tarda induced by estrogens. Arch Dermatol. (Three cases of men given diethylstilbestrol for prostate cancer who developed porphyria cutanea tarda 8-48 months later).
Holzbach RT, Sanders JH. (1965). Recurrent intrahepatic cholestasis of pregnancy: observations on pathogenesis. JAMA. (32 year old woman developed severe, generalized pruritus in last trimester of 3 pregnancies, followed by mild jaundice during fourth pregnancy [bilirubin 4.0 mg/dL, AST 92 U/L, Alk P 3 times ULN] and then redeveloped symptoms and laboratory test abnormalities 1-2 weeks after starting OCCs; mother and sister had similar symptoms during pregnancies).
Perlroth MG, Marver HS, Tschudy DP. (1965). Oral contraceptive agents and the management of acute intermittent porphyria. JAMA. (Report of three women with cyclic premenstrual exacerbations of porphyria in whom OCCs appeared to control symptoms).
von Oldershausen H-F, Eggstein M, Dold U, Knörr K. (1965). Dtsch Med Wochenschr. (31 year old woman developed pruritus 3 weeks and jaundice 5 weeks after starting OCCs [bilirubin 6.9 mg/dL], resolving slowly after stopping [>3 months] despite corticosteroid therapy).
von Oldershausen HF, Eggstein M, Dold U, Knörr K. (1966). Intrahepatic cholestasis with jaundice after taking contraceptive steroids. Ger Med Mon. (English translation of von Oldershausen [1965] of 31 year old woman with cholestasis due to OCCs).
Schaffner F. (1966). The effect of oral contraceptives on the liver. JAMA. (Review of literature on effects of OCCs on the liver and recommendations on their avoidance in women with history of jaundice of pregnancy, primary biliary cirrhosis and constitutional hyperbilirubinemia).
Ecker JA, McKittrick JE, Failing RM. (1966). Thrombosis of the hepatic veins. The Budd-Chiari syndrome a possible link between oral contraceptives and thrombosis formation. Am J Gastroenterol. (23 year old woman developed nausea and acute abdominal pain within weeks of starting OCCs with progression to massive ascites and hepatic failure; hepatic vein thrombosis found on autopsy).
Orellana-Alcalde JM, Dominguez JP. (1966). Jaundice and oral contraceptive drugs. Lancet. (Over 50 women with jaundice on OCCs seen over a two year period in Santiago, Chile; geographic distribution similar to intrahepatic cholestasis of pregnancy; estrogen usually ethinylestradiol 0.05 mg or mestranol 0.15 mg daily; 17 of 42 had previous history of cholestasis during pregnancy; onset usually with first cycle; bilirubin 1.7-19.3 mg/dL, Alk P mildly elevated and ALT raised in two-thirds, some above 300 U/L; positive rechallenge in 6).
Thulin KE, Nermark J. (1966). Seven cases of jaundice in women taking oral contraceptive, Anovlar. Br Med J. (Six women on OCC [Anovlar] seen with jaundice in two month period; ages 19-37 years on OCCs for unknown duration [bilirubin 3.0-8.1 mg/dL, ALT 115-1600 U/L, Alk P 1-2 times ULN]; one had history of pruritus of pregnancy).
Copeman PW, Cripps DJ, Summerly R. (1966). Cutaneous hepatic porphyria and oestrogens. Br Med J. (Two men with prostate cancer treated with estrogen therapy developed cutaneous manifestations of porphyria, but with little change in serum, urine or fecal porphyrin excretion).
Card IR, Sneddon IB, Talbot CH. (1966). Oral contraceptives and jaundice. Br Med J. (34 year old woman on OCCs for 2 years developed severe pruritus without jaundice [bilirubin 1.6-2.4 mg/dL, Alk P 1.5-2.5 times ULN], with resolution on stopping OCCs; had history of pruritus of pregnancy).
Kreek MJ, Weser E, Sleisenger MH, Jefferies GH. (1967). Idiopathic cholestasis of pregnancy: the response to challenge with the synthetic estrogen, ethinyl estradiol. N Engl J Med. (7 women with a history of pruritus or jaundice of pregnancy and 6 controls were treated with ethinyl estradiol [0.5 to 1.5 mg daily] for up to two weeks; estrogens triggered symptoms of pruritus in most women with a history of cholestasis of pregnancy, marked rise in BSP retention and jaundice [bilirubin 2.4 mg/dL] in one; no change in the controls).
Sterup K, Mosbech J. (1967). Budd-Chiari syndrome after taking oral contraceptives. BMJ. (28 year old woman taking OCCs for 12-18 months developed nausea and abdominal distention, with progressive ascites and variceal hemorrhage; autopsy showed hepatic vein thrombosis).
Medical Research Council. (1967). Risk of thromboembolic disease in women taking oral contraceptives. Br Med J. (Two small case controlled studies in general practice population found link between OCCs and venous thrombosis and pulmonary embolus, but not coronary thrombosis).
Grayson MJ, Reilly MCT. (1968). Budd-Chiari syndrome after oral contraceptives. BMJ. (37 year old woman on OCCs for a year developed pain and abdominal distension with acute Budd-Chiari syndrome and death).
Clubb AW, Giles C. (1968). Budd-Chiari syndrome in women taking oral contraceptives. Br Med J. (40 year old woman on OCCs for 2 years underwent surgery for uterine fibroids and was found to have an enlarged liver developing progressive ascites in postoperative period leading to hepatic failure and death; autopsy showed thrombosis in hepatic veins).
Rothwell-Jackson RL. (1968). Budd Chiari syndrome after oral contraceptives. Br Med J. (24 year old woman developed Budd-Chiari syndrome 4 months after starting OCCs, with progressive course and death, autopsy showing hepatic vein thrombosis).
Somayaji BN, Eeles GH, Paton A, Parker RGF. (1968). Budd-Chiari syndrome after oral contraceptives. Br Med J. (39 year old woman developed Budd Chiari syndrome after taking OCCs for 2.5 years; improved without surgery on stopping OCCs).
Somayaji BN, Paton A, Price JH, Harris AW, Flewett TH. (1968). Norethisterone jaundice in two sisters. Br Med J. (Two sisters developed jaundice and pruritus after taking OCCs or estrogens for 18 and 10 days [bilirubin 6.7 and 12.8 mg/dL, ALT 30 and 16 U/L, Alk P ~3 times ULN], with slow recovery on stopping pill; one had history of pruritus of pregnancy).
Chamberlain DW, Walter JB. (1969). The relationship of Budd-Chiari syndrome to oral contraceptives and trauma. Can Med Assoc J. (37 year old on OCCs for two years developed acute Budd-Chiari syndrome after a motor vehicle accident and abdominal trauma).
Irey NS, Manion WC, Taylor HB. (1970). Vascular lesions in women taking oral contraceptives. Arch Pathol. (Analysis of arteries and veins from tissue specimens from 20 women who developed thromboembolism during OCC therapy [5 weeks to 13 months]; one had Budd Chiari syndrome, found locally formed thrombi rather than thromboembolus, changes in walls at site of thrombi suggesting that these were primary).
Adlercreutz H, Tenhunen R. (1970). Some aspects of the interaction between natural and synthetic female sex hormones and the liver. Am J Med. (Review of effects of estrogens on hepatic function in relationship to cholestasis of pregnancy and cholestasis induced by estrogens and OCCs).
Kositchek RJ, Cullen RA. (1970). Hemangiomatosis of the liver with thrombosis following use of an oral contraceptive. Calif Med. (36 year old woman on cyclic estrogen therapy for menorrhagia for 6 months developed hepatic mass, wedge biopsy showing hemangiomatosis, stable upon stopping therapy but few details given).
Rowley PT, Kurnick J, Cheville R. (1970). Hereditary haemorrhagic telangiectasia: aggravation by oral contraceptives. Lancet. (Reports of three women who had worsening problems with telangiectasia after starting OCCs including increase in size and more frequent bleeding).
Harris PW. (1970). Hereditary haemorrhagic telangiectasia and oral contraceptives. Lancet. (Suggests that higher doses of estrogens are needed to control epistaxis and that lower doses might worsen telangiectasia).
Blackburn EK. (1970). Hereditary haemorrhagic telangiectasia and oral contraceptives. Lancet. (Comments on acne being worsened by some estrogen preparations).
Harrison DF. (1970). Hereditary haemorrhagic telangiectasia and oral contraceptives. Lancet. (Unlike Rowley et al, this investigator found improvement in bleeding episodes in patients with hereditary telangiectasia with estrogen or OCC therapy).
Hoyumpa AM, Schiff L, Helfman EL. (1971). Budd-Chiari syndrome in women taking oral contraceptives. Am J Med. (Two women developed Budd Chiari syndrome 3 weeks and 8 years after starting OCCs; one survived with diuretic therapy, the other died).
Dooner HP, Hoyl C, Aliaga C, Parada J. (1971). Jaundice and oral contraceptives. Acta Hepatosplenol. (Seven women who developed jaundice on OCCs, cholestatic in 6, details given in two patients).
Kontturi M, Sotaniemi E, Ahlgvist J. (1972). Liver damage and estrogen therapy of prostatic cancer: case report. Scand J Urol Nephrol. (Among 62 men with prostate cancer treated with diethylstilbestrol, 1 developed jaundice 40 days after starting [bilirubin 6.9 mg/dL, but normal ALT and Alk P], resolved on stopping, but later found to have cirrhosis).
Metreau JM, Dhumeaux D, Berthelot P. (1972). Oral contraceptives and the liver. Digestion. (Review of effects of OCCs on the liver; over 300 cases of jaundice due to OCCs have been reported with higher frequency in Chile and Scandinavia [1:4000 cases vs 1:10,000 elsewhere); higher rate with early OCCs such as Lyndiol, Anovlar and Enovid compared to later, lower dose preparations]).
Johnson FL, Lerner KG, Siegel M, Feagler JR, Majerus PW, Hartmann JR, Thomas ED. (1972). Association of androgenic-anabolic steroid therapy with the development of hepatocellular carcinoma. Lancet. (Description of 4 cases of hepatocellular carcinoma related to C17-alkylated anabolic steroids given for aplastic anemia or Fanconi syndrome, 2 females and 2 males, ages 5 to 27 years taking drugs for 1-7 years; regression of tumor in one after withdrawal but all died within one year).
Cohen L, Lewis C, Arias IM. (1972). Pregnancy, oral contraceptives, and chronic familial jaundice with predominantly conjugated hyperbilirubinemia(Dubin-Johnson syndrome). Gastroenterology. (Among 101 patients seen for jaundice during pregnancy or OCC use, 27 had Dubin-Johnson syndrome, marked by normal serum enzymes and bile acids; onset of jaundice during first 3 cycles of OCCs or late in pregnancy, rapid reversal with stopping or delivery; family studies suggested autosomal recessive inheritance; liver biopsies were black with pericanalicular black pigment).
Rencoret R, Aste H. (1973). Jaundice during pregnancy. Med J Aust. (32 cases of jaundice during pregnancy, 0.43% of all pregnancies [Chile]; usually arising in 3rd trimester, 50% recurrence after initial episode; pruritus followed in 2-3 weeks by jaundice, but bilirubin rarely above 5.0 mg/dL, Alk P elevated 1-6 times ULN and ALT elevations up to 176 U/L, often leading to prematurity, resolves rapidly with delivery; no maternal deaths).
Baum JK, Brookstein JJ, Holtz F, Klein EW. (1973). Possible association between benign hepatomas and oral contraceptives. Lancet. (Seven cases of hepatic adenoma in woman on OCCs for 0.5-7 years, ages 25 to 39 years, 5 with rupture, one fatal).
Contostavlos DL. (1973). Benign hepatomas and oral contraceptives. Lancet. (37 year old woman on OCCs for many years developed acute epigastric pain and died suddenly, autopsy showing large adenoma).
Boston Collaborative Drug Surveillance Programme. (1973). Oral contraceptives and venous thromboembolic disease, surgically confirmed gallbladder disease, and breast tumours. Lancet. (Hospital based survey of women ages 20 to 44 years found higher rates of OCC use among those with diagnosis of venous thromboembolism [72% vs 20% in controls] and gallbladder disease [31% vs 20%], but not breast tumors).
Boston Collaborative Drug Surveillance Program. (1974). Surgically confirmed gallbladder disease, venous-thromboembolism and breast tumors in relation to postmenopausal estrogen therapy. N Engl J Med. (Hospital based survey of 5339 postmenopausal women, ages 45 to 69 years, found higher rate of gall bladder disease in women on estrogens; relative risk of 2.5, but no association of estrogen use with thromboembolism or breast cancer).
Berg JW, Ketalaar RJ, Rose EF, Vernon RG. (1974). Letter. Hepatomas and oral contraceptives. Lancet. (During 3 year period, 4 women with hepatic adenomas were entered in an Iowa State registry, ages 23 to 32 years, 3 on OCCs and one pregnant; no cases in previous 35 years).
O'Sullivan JP, Wilding RP. (1974). Liver hamartomas in patients on oral contraceptives. Br Med J. (3 cases of liver tumors arising in 34, 35 and 51 year old women on OCCs for 4-8 years, referred to as hamartomas, but later said to be more likely adenomas).
Thalassinos NC, Lymberatos C, Hadjioannou J, Gardikas C. (1974). Liver-cell carcinoma after long-term oestrogen-like drugs. Lancet. (30 year old woman treated with estrogens for infertility developed 5 cm hepatocellular carcinoma shortly after delivery).
Kelso DR. (1974). Benign hepatomas and oral contraceptives. Lancet. (36 year old woman on OCCs for 5 years had acute hemoperitoneum from large hepatic adenoma and died).
Meyer P, Livolsi VA, Cornog JL. (1974). Hepatoblastoma associated with an oral contraceptive. Lancet. (19 year old woman on OCCs for 9 months developed fever and abdominal pain and found to have a 17 cm locally invasive hepatoblastoma).
Tountas C, Paraskevas G, Deligeorgi H. (1974). Benign hepatoma and oral contraceptives. Lancet. (30 year old woman on OCCs for 3 years had successful resection of hepatic adenoma).
Dalén E, Westerholm B. (1974). Occurrence of hepatic impairment in women jaundiced by oral contraceptives and in their mothers and sisters. Acta Med Scand. (Questionnaire from 141 women with OCC associated jaundice and 210 controls on OCCs without problems; 47% of patients had pruritus and 6% jaundice during pregnancy compared to 11% and 0 in controls; also higher rate of gallstones [20% vs 4%], and pruritus/jaundice during pregnancy [15% vs 1%] among siblings of patients compared to controls).
Drill VA. (1974). Benign cholestatic jaundice of pregnancy and benign cholestatic jaundice from oral contraceptives. Am J Obstet Gynecol. (Review of clinical presentation and pathogenesis of cholestasis of pregnancy and OCCs).
Morley JE, Myers JB, Sack PS, Kalk F, Epstein EE, Lannon J. (1974). Enlargement of cavernous haemangioma associated with exogenous administration of oestrogens. S Afr Med J. (57 year old woman developed enlarging hepatic mass on estrogens; 950 gram cavernous hemangioma).
Frederick WC, Howard RG, Spatola S. (1974). Spontaneous rupture of the liver in a patient using contraceptive pills. Arch Surg. (28 year old woman on OCCs for 14 months presented with spontaneous rupture of liver; resected lobe showed hepatic vein thrombosis without tumor).
Knapp WA, Ruebner BH. (1974). Hepatomas and oral contraceptives. Lancet. (33 year old woman on OCCs for several years presented with acute abdomen and was found to have large adenoma, died postoperatively).
Horvath E, Kovacs K, Ross RC. (1974). Letter: Benign hepatoma in a young woman on contraceptive steroids. Lancet. (28 year old on OCCs for 7 years had adenoma, on electron microscopy cells had crystalloid inclusions in mitochondria).
Albritton DR, Tompkins RK, Longmire WP. (1974). Hepatic cell adenoma: a report of four cases. Ann Surg. (Four cases of hepatic adenoma undergoing resection; no mention of OCCs).
Mays ET, Christopherson WM, Burrows GH. (1974). Focal nodular hyperplasia of the liver – possible relationship to oral contraceptives. Am J Clin Pathol. (Three women on OCCs for 4-7 years found to have large hepatic masses after presenting with pain or hemoperitoneum; appeared to be focal nodular hyperplasia rather than adenomas).
Winkler K, Poulsen H. (1975). Liver disease with periportal sinusoidal dilatation. Scand J Gastroenterol. (Four women on OCCs who underwent liver biopsy for different indications were found to have sinusoidal dilatation in periportal [zone 1] areas).
Christopherson WM, Mays ET, Barrows GH. (1975). Liver tumors in women on contraceptive steroids. Obstet Gynecol. (Pathology report on 13 cases of liver tumors in women on OCCs including 8 with focal nodular hyperplasia, 3 hamartoma, 1 adenoma and 1 carcinoma).
Davis M, Portmann B, Searle M, Wright R, Williams R. (1975). Histological evidence of carcinoma in a hepatic tumour associated with oral contraceptives. Br Med J. (21 year old woman on OCCs for 2 years found to have 820 g hepatic mass which had histological features of focal nodular hyperplasia and hepatocellular carcinoma; only short term follow up given).
Antoniades K, Brooks CE. (1975). Hemoperitoneum from liver cell adenoma in a patient on oral contraceptives. Surgery. (30 year old woman had spontaneous rupture of 6.5 cm adenoma 5 weeks after third pregnancy; history of OCC use for 4 years).
Antoniades K, Campbell WN, Hecksher RH, Kessler WB, McCarthy GE. (1975). Liver cell adenoma and oral contraceptives: double tumor development. JAMA. (32 year old woman on OCCs for 6 years presented with abdominal pain and found to have two hepatic masses, 14 and 7.5 cm hepatic adenomas).
Ameriks JA, Thompson NW, Frey CF, et al. (1975). Hepatic cell adenomas. Spontaneous liver rupture and oral contraceptives. Arch Surg. (Review of 8 cases of hepatic adenoma seen in 5 years at one center; all were women, ages 25 to 44 years taking OCCs for 6 months to 9 years).
Stenwig AE, Solgaard T. (1975). Ruptured benign hepatoma associated with an oral contraceptive. A case report. Virchows Arch A Pathol Anat Histol. (Rupture of hepatic adenoma late in pregnancy of a woman who had been on OCCs for 8 years).
Grabowski M, Stenram U, Bergvist A. (1975). Focal nodular hyperplasia of the liver, benign hepatomas, oral contraceptives and other drugs affecting the liver. Acta Pathol Microbiol Scand A. (Retrospective review of pathology files from two hospitals identified 18 cases of focal nodular hyperplasia and 2 cases of adenoma in women; half were taking OCCs).
Langlands AO, Martin WM. (1975). Jaundice associated with norethisterone-acetate treatment of breast cancer. Lancet. (107 patients with breast cancer were treated with progesterone derivative; 6 developed jaundice within 4 months with elevations in ALT [192-287 U/L] and Alk P [1-5 times ULN] and mild jaundice that resolved with stopping).
Stauffer JQ, Lapinski MW, Honold DJ, Myers JK. (1975). Focal nodular hyperplasia of the liver and intrahepatic hemorrhage in young women on oral contraceptives. Ann Intern Med. (Three women presenting with pain and liver masses on long term OCCs [6-7 years] found to have focal nodular hyperplasia on resection).
Knowles DM, Wolff M. (1975). Systemic contraceptives and the liver. Ann Intern Med. (Letter to editor in response to Stauffer [1975] stressing the importance but difficulty in separating adenomas from focal nodular hyperplasia).
Haberman HF, Rosenberg F, Menon IA. (1975). Porphyria cutanea tarda: comparison of cases precipitated by alcohol and estrogens. Can Med Assoc J. (7 patients with porphyria cutanea tarda [PCT] precipitated by alcohol were compared to 9 patients with PCT precipitated by estrogens; similar clinical features; estrogens taken for 7 months to 14 years; some, but not all had AST elevations or high iron indices; stopping estrogens reversed symptoms in only one patient; all responded to phlebotomy).
Glassberg AB, Rosenbaum EH. (1976). Letter: Oral contraceptives and malignant hepatoma. Lancet. (31 year old woman on OCCs for 11 years was found to have a large hepatic mass and secondary lesions shown histologically to be hepatocellular carcinoma; no details of follow up given).
Hilliard JL, Graham DY, Spjut HJ. (1976). Hepatic adenoma: a possible complication of oral contraceptive therapy. South Med J. (Three cases of hepatic adenomas in women, two on OCCs for 1.2 and 4 years).
Kalra TM, Mangla JC, DePapp EW. (1976). Benign hepatic tumors and oral contraceptive pills. Am J Med. (10 year retrospective review of records from 5 hospitals; found 7 adenomas, 5 in young women [ages 29 to 40 years] on OCCs and 2 cases of peliosis in 8 and 64 year olds, both with aplastic anemia on androgenic steroids).
Lansing PB, McQuitty JT, Bradburn DM. (1976). Benign liver tumors: what is their relationship to oral contraceptives?. Am Surg. (Between 1952-75, authors identified 3 cases of adenoma and 5 of focal nodular hyperplasia, 7 in women, all survived after resection; 5 had taken OCCs).
Tigano F, Ferlazzo B, Barrile A. (1976). Oral contraceptives and malignant hepatoma. Lancet. (22 year old woman on OCCs for 2 years developed hepatocellular carcinoma and died; viral markers not reported).
McAvoy JM, Tompkins RK, Longmire WP. (1976). Benign hepatic tumors and their association with oral contraceptives. Arch Surg. (Two women on OCCs for 15 and 9 years presented with large hepatic masses, found to be adenoma on resection: review of literature).
Andersen PH, Packer JT. (1976). Hepatic adenoma: observations after estrogen withdrawal. Arch Surg. (24 year old woman on OCCs for 20 months presented with hepatic rupture and biopsy showed adenoma, but tumor incompletely resected; OCCs stopped and tumor decreased in size, but ultimately required resection 18 months later).
Brander WL, Vosnides G, Ogg CS, West IE. (1976). Multiple hepatocellular tumors in a patient treated with oral contraceptives. Virchows Arch A Pathol Anat Histol. (24 year old woman with chronic renal failure developed large liver and spontaneous rupture; autopsy showed 5 kg liver with multiple adenomas).
Edmondson HA, Reynolds TB, Henderson B, Benton B. (1976). Liver cell adenomas associated with use of oral contraceptives. N Engl J Med. (Analysis of 42 women with hepatic adenomas and matched controls; OCC use was common [85 vs 70%] and used for longer in those with adenomas [80 vs 38 months] and higher mestranol vs ethinyl estradiol use).
Mays ET, Christopherson WM, Mahr MM, Williams HC. (1976). Hepatic changes in young women ingesting contraceptive steroids: hepatic hemorrhage and primary tumors. JAMA. (Review of 13 women presenting with liver tumors on OCCs seen between 1968-74; none had cirrhosis; 9 tumors were benign [mostly focal nodular hyperplasia; all alive] and 4 malignant [hepatocellular carcinoma; 3 died]; 6 presented with rupture, one tumor recurred in woman who continued OCC use).
Ross D, Pina J, Mirza M, Galvan A, Ponce L. (1976). Letter: Regression of focal nodular hyperplasia after discontinuation of oral contraceptives. Ann Intern Med. (25 year old woman on OCCs for 6 years presented with several hepatic masses, one resected showed probable adenoma, the other regressed in size during follow up off of OCCs).
Goldfarb S. (1976). Sex hormones and hepatic neoplasia. Cancer Res. (Review of literature and 6 cases of liver tumors related to estrogens and OCCs: among 40 cases in the literature, 25 were called adenoma, 13 focal nodular hyperplasia, 3 hamartomas, 3 carcinoma and 1 hepatoblastoma; a major problem was lack of consistency in histologic criteria for diagnosis).
Alpert LI. (1976). Veno-occlusive disease of the liver associated with oral contraceptives. Case report and review of literature. Hum Pathol. (36 year old woman on OCCs for 4 years developed ascites, esophageal varices and progressive hepatic failure; autopsy showed hepatic vein thrombosis and obliteration of hepatic veins suggestive of veno-occlusive disease).
de Pagter AG, van Berge Henegouwen GP, ten Bokkel Huinink JA, Brandt KH. (1976). Familial benign recurrent intrahepatic cholestasis. Interrelation with intrahepatic cholestasis of pregnancy and from oral contraceptives?. Gastroenterology. (Study of a family with 4 members with benign recurrent intrahepatic cholestasis [BRIC], 9 with cholestasis of pregnancy and two with cholestasis on OCCs; one BRIC patient had recurrent episodes of cholestasis during pregnancies; suggesting shared pathogenesis of these three cholestatic syndromes).
Medline A, Ptak T, Gryfe A, Blenkinsop B. (1976). Pruritus of pregnancy and jaundice induced by oral contraceptives. Am J Gastroenterol. (18 year old woman developed jaundice 1 month after starting OCCs and then pruritus of pregnancy in third trimester; jaundice recurrence on restarting OCCs which were continued until bilirubin reached 37 mg/dL, AST 114 U/L, Alk P 306 U/L, resolving on stopping).
Edmondson HA, Reynolds TB, Henderson B, Benton B. (1977). Regression of liver cell adenomas associated with oral contraceptives. Ann Intern Med. (Three women on OCCs for 4-13 years found to have multiple or unresectable hepatic adenomas with regression after stopping).
Leissner KH, Wedel H, Scherstein T. (1977). Comparison between the use of oral contraceptives and the incidence of surgically confirmed gallstone disease. Scand J Gastroenterol. (Analysis of cholecystectomy rates in Sweden from 1961-71; there was an increase in rates in women who were 20-54 years old, suggestive of an effect of introduction of OCCs in early 1960s).
Christopherson WM, Mays ET. (1977). Liver tumors and contraceptive steroids: experience with the first one hundred registry patients. J Natl Cancer Inst. (Analysis of first 100 patients in a registry of liver tumors in women found 40 adenomas, 44 focal nodular hyperplasias, 13 liver cancers and 4 unclassified tumors, mean age 30 years [14 to 47 years], only 4 were never on OCCs, pregnant or on estrogens [4-156 months]; presenting as hemoperitoneum [26%], pain [32%], mass [19%] or incidental finding [20%]).
Nissen ED, Kent DR, Nissen SE. (1977). Etiologic factors in the pathogenesis of liver tumors associated with oral contraceptives. Am J Obstet Gynecol. (Registry of liver tumors and review of literature identified 71 cases of benign liver tumors associated with OCCs).
Aldinger K, Ben-Manachem Y, Whalen G. (1977). Focal nodular hyperplasia of the liver associated with high-dosage estrogens. Arch Intern Med. (32 year old woman on estrogens after oophorectomy developed enlarging hepatic mass; on resection 4 years later it was at 10 cm focal nodular hyperplasia; on continuing estrogens she developed further hepatic masses than regressed when estrogens were stopped).
Klatskin G. (1977). Hepatic tumors. Possible relationship to use of oral contraceptives. Gastroenterology. (Between 1973-75, reports of 237 hepatic tumors in women on OCCs; 44% adenomas, 35% focal nodular hyperplasia, 8% hepatocellular carcinoma; among benign tumors, 93% survival, recurrence only in patients who continued OCCs; among malignant tumors, survival ~50%, recurrence uncommon; discusses difficulty in diagnosis of adenoma vs focal nodular hyperplasia even with strict criteria).
Vana J, Murphy GP, Aronoff BL, Baker HW. (1977). Study of association between liver tumors and oral contraceptive use. JAMA. (American College of Surgeon’s survey for 1970-75 identified 212 benign tumors in women; 96 adenomas and 58 focal nodular hyperplasia; OCC use reported in 74% of women with both types of tumors, but no evidence of dose-response; increase in yearly numbers of benign tumors between 1970 [n=22] and 1975 [n=47]).
Blayney AW, O’Callaghan T, MacErlean DP, O’Connell TC. (1977). Fatal outcome of an hepatic adenoma follow short term oral contraceptive use. Ir Med J. (30 year old on OCCs for 18 months presented with intrahepatic bleed due to 12 cm hepatic adenoma in normal liver; sudden death).
Kay S. (1977). Nine-year follow up of a case of benign liver cell adenoma related to oral contraceptives. Cancer. (26 year old woman on OCC developed adenoma that was successfully resected, recurrence at 3 years during continuation of OCCs and regression over 6 years with stopping).
Anonymous. (1977). Liver tumours and the pill. Br Med J. (Editorial on association of OCC and liver tumors: over 200 cases reported usually in long-term users of OCC with no accompanying liver disease).
Barrows GH, Christopherson WM, Drill VA. (1977). Liver lesions and oral contraceptive steroids. J Toxicol Environ Health. (No increase in hepatic tumors in two strains of mice given OCCs).
Wu SM, Spurny OM, Klotz AP. (1977). Budd-Chiari syndrome after taking oral contraceptives. A case report and review of 14 reported cases. Am J Dig Dis. (24 year old woman on OCCs for 4 years presented with abdominal pain and ascites and found to have Budd Chiari syndrome).
Pryor AC, Cohen RJ, Goldman RL. (1977). Hepatocellular carcinoma in a woman on long-term oral contraceptives. Cancer. (32 year old woman on OCCs for 12 years presented with large hepatocellular carcinoma and died 1.5 years later of disease progression).
Chan CK, Detmer DE. (1977). Proper management of hepatic adenoma associated with oral contraceptives. Surg Gynecol Obstet. (In instances without rupture, authors recommend stopping OCCs and observation, reserving resection for large tumors to be done by experienced surgeons only).
Fechner RE. (1977). Benign hepatic lesions and orally administered contraceptives: a report of severe cases and a critical analysis of the literature. Hum Pathol. (Case series and clinical description of 12 young women with benign hepatic tumors; 6 adenomas [5 on OCCs] and 6 focal nodular hyperplasia [2 on OCCs], and extensive review of the literature).
Jick H, Herman R. (1978). Oral contraceptive-induced benign liver tumors-the magnitude of the problem. JAMA. (From 2 retrospective studies, estimates were made that 100-140 U.S. women on OCCs developed hepatic tumors each year since 1970; or 1:80,000 users).
Kent DR, Nissen ED, Nissen SE, Ziehm DJ. (1978). Effect of pregnancy on liver tumor associated with oral contraceptives. Obstet Gynecol. (Among 80 cases of liver tumors in OCC users in a registry, 4 cases had complications of adenomas during pregnancy, 2 presenting with rupture and 2 with enlarging mass and pain, usually during last trimester, suggesting that pregnancy is associated with tumor growth).
Trias R, Rius X, Autonell J, Algaba F. (1978). Hepatocarcinoma and oral contraceptives. Lancet. (28 year old woman on OCCs for 13 months presented with 18 cm hepatocellular carcinoma with normal remaining liver).
Taxy JB. (1978). Peliosis. A morphologic curiosity becomes an iatrogenic problem. Hum Pathol. (Five patients presenting with peliosis hepatis [4 with splenic involvement], all had received androgenic steroids or chemotherapy for lymphoma or myeloproliferative diseases).
Nime F, Pickren JW, Vana J, Aronoff BL, Baker HW, Murphy GP. (1979). The histology of liver tumors in oral contraceptive users during a national survey by the American College of Surgeons Commission on Cancer. Cancer. (Analysis of 94 submitted slides from liver tumors; 39% adenomas, 56% focal nodular hyperplasia [FNH]; all reported hamartomas were considered to be FNH; adenomas were larger than FNH and found only in OCC users, whereas FNH cases in OCC users had more vascular changes including peliosis).
Rooks JB, Ory HW, Ishak KG, Straus LT, Greenspan JR, Hill AP, Tyler CW, Cooperative Liver Tumor Study Group. (1979). Epidemiology of hepatocellular adenoma. The role of oral contraceptive use. JAMA. (Case control study of 79 young women with hepatic adenomas from the files of the Armed Forces Institute of Pathology compared to 299 controls, found increasing relative risk with long term OCC use from 1 ≤12 months to 129 for greater than 5 years; rate estimate of 3.4/100,000 patient years).
Pollak H. (1979). MMW Munch Med Wochenschr. (34 year old woman on OCCs for 10 years developed sudden onset of right upper quadrant pain and shock and was found to have ruptured adenoma).
Sabriá Leal M, Mateu Ratera M, Canals Cadafalch J, Blanch Mortes MD, Munuera Gifre E. (1979). Med Clin (Barc). (Two women, ages 30 and 35 years, on OCCs for 4 and 5 years, presented with pain and hepatic mass, found to have large hepatic adenomas).
Ham JM, Fracs F, Pirola RC, Couch RL. (1980). Hemangioendothelial sarcoma of the liver associated with long-term estrogen therapy in a man. Dig Dis Sci. (81 year old man with prostate cancer treated with stilbestrol for 9 years presented with pain and jaundice with bilirubin 4.1 mg/dL, mass on liver scan and autopsy showing large tumor consisting of large vascular spaces “hemangioenothelial sarcoma”).
Bartók I, Decastello A, Csikós F, Nagy I. (1980). Focal nodular hyperplasia of the liver and hepatic cell adenoma in women on oral contraceptives. Hepatogastroenterology. (Two women, ages 34 and 41 years, had onset of abdominal pain after 5 and 10 years of OCC use and found to have hepatic masses; one a 6 cm mass of focal nodular hyperplasia; the second a 19 cm adenoma; both successfully resected).
Neuberger J, Portmann B, Nunnerley HB, Laws JW, Davis M, Williams R. (1980). Oral-contraceptive-associated liver tumours: occurrence of malignancy and difficulties in diagnosis. Lancet. (Experience at King’s College Liver Unit, London between 1970-79; 10 women ages 12 to 42 years were found with hepatic tumors who had been on OCCs for 4-12 years, 7 were hepatocellular carcinoma; usually had Alk P elevations, minimal increases in AST; alpha-fetoprotein was always normal; 4 died of metastatic disease).
Littlewood ER, Harrison IG, Murray-Lyon IM, Paradinas FJ. (1980). Cholangio-carcinoma and oral contraceptives. Lancet. (21 year old on OCCs for 5 years found to have cholangiocarcinoma; HBsAg and alpha-fetoprotein negative; no follow up given).
Camilleri M, Schafler K, Chadwich VS, Hodgson JH, Weinbren K. (1981). Periportal sinusoidal dilatation, inflammatory bowel disease, and the contraceptive pill. Gastroenterology. (Two women, ages 19 and 28 year old, developed fatigue, diarrhea and weight loss 1.5 and 7 years after starting OCCs [bilirubin normal, AST 60 U/L and normal, Alk P 186 and 204 U/L], with hepatomegaly and liver biopsy showing periportal peliosis; symptoms [including diarrhea] and liver test abnormalities resolving within 2-4 weeks on stopping OCCs).
Tesluk H, Lawrie J. (1981). Hepatocellular adenoma: its transformation to carcinoma in a user of oral contraceptives. Arch Pathol Lab Med. (34 year old woman on OCCs for 5 years presented with 14 cm adenoma which regressed in size with stopping; 3 years later the tumor began to grow and she underwent resection which showed hepatocellular carcinoma; patient died due to surgical complications).
Christensen SE, Andersen VR, Vilstrup H. (1981). A case of hepatoma in pregnancy associated with earlier oral contraception: a case report. Acta Obstet Gynecol Scand. (45 year old woman developed hepatocellular carcinoma in last trimester of pregnancy; had taken OCCs for 5 years, 8 years before presentation).
Penkava RR, Rothenberg J. (1981). Spontaneous resolution of oral contraceptive-associated liver tumor. J Comput Assist Tomogr. (55 year old woman presented with rupture of hepatic adenoma after 10 years of OCC use, repeat CT scans in follow up showed shrinkage after stopping).
Monroe PS, Roddell RH, Siegler M, Baker AL. (1981). Hepatic angiosarcoma: possible relationship to oral contraceptive ingestion. JAMA. (32 year old woman on OCCs for 8 years developed multiple hepatic masses; surgery showed angiosarcoma [factor VIII positive]; tumor remained stable after stopping OCCs).
Porter JB, Jick H, Ylvisaker JT. (1981). Malignant liver tumor associated with oral contraceptive use. Pharmacotherapy. (38 year old woman on OCCs for 10 years presented with abdominal mass found on autopsy to be cholangiocarcinoma).
Capron J-P, Lemay J-L, Muir J-F, Dupas JL, Lebrec D, Gineston JL. (1981). Portal vein thrombosis and fatal pulmonary thromboembolism associated with oral contraceptive treatment. J Clin Gastroenterol. (33 year old woman on OCCs for 8 years found to have portal vein thrombosis and varices; died of multiple pulmonary emboli; likely had hypercoagulable state).
Balázs M, Kovách G, Winkler G, Jánossy J. (1981). Dtsch Med Wochenschr.
Steinbrecher UP, Lisbona R, Huang SN, Mishkin Sl. (1981). Complete regression of hepatocellular adenoma after withdrawal of oral contraceptive use. Dig Dis Sci. (28 year old woman on OCCs for 10 years presented with hepatic adenoma which regressed within 12 months of stopping: Case 3).
Thung SN, Gerber MA. (1981). Precursor stage of hepatocellular neoplasm following long exposure to orally administered contraceptives. Hum Pathol. (32 year old woman with Crohn's disease on OCCs for 10 years found to have Alk P 600 U/L, ALT 25 U/L, bilirubin 1.0 mg/dL and biopsy showing peliosis, increased reticulum and thick walled arteries and fibrosis in portal areas).
Ishak KG. (1981). Hepatic lesions caused by anabolic and contraceptive steroids. Semin Liver Dis. (Review of histologic effects of male and female sex hormones on the liver including biochemical changes, subcellular alternations, cholestasis, vascular disorders, hyperplasia, neoplasia and miscellaneous).
Shi EC, Fischer A, Crouch R, Ham JM. (1981). Possible association of angiosarcoma with oral contraceptive agents. Med J Aust. (42 year old woman who had taken OCCs for 10 years presented one year after stopping with unresectable hepatic mass; 15 cm angiosarcoma on autopsy).
Mettlin C, Nachimuthu N. (1981). Studies on the role of oral contraceptive use in the etiology of benign and malignant liver tumors. J Surg Oncol. (Chronological review of the literature linking OCCs and hepatic tumors; case-control studies have demonstrated a clear relationship of OCCs and hepatic adenomas, associated with longer duration of use and perhaps type of OCC; OCCs may also predispose to rupture and perhaps promote growth of unrelated benign lesions; their oncogenic potential requires further investigation).
Lockhat D, Katz SS, Lisbona R, Mishkin S. (1981). Oral contraceptives and liver disease. Can Med Assoc J. (19 year old woman on OCCs for 2.5 years developed abdominal pain and bloating [bilirubin 1.8 mg/dL, Alk P 114 U/L, ALT 35 U/L]; fluid in peritoneum and biopsy showed Budd-Chiari syndrome, with subsequent improvement after porto-caval shunt).
Schonberg LA. (1982). Peliosis hepatis and oral contraceptives. A case report. J Reprod Med. (36 year old woman developed tender liver with normal serum enzymes; laparotomy showed ascites and hepatomegaly, while liver biopsy showed peliosis hepatis; OCCs stopped, but no follow up given).
Royal College of General Practitioners Oral Contraception Study. (1982). Oral contraceptives and gallbladder disease. Lancet. (Analysis of frequency of gallbladder disease among OCC users and matched controls showed increased risk with OCC use in early years that was later followed by decreased risk, making the overall association questionable; “it is unlikely that all the previous studies were incorrect”).
Helling TS, Wood WG. (1982). Oral contraceptives and cancer of the liver: a review with two additional cases. Am J Gastroenterol. (21 and 33 year old women on OCCs for 2 and 15 years presented with abdominal pain and found to have hepatocellular carcinoma without cirrhosis, both dying within a year).
Goodman ZD, Ishak KG. (1982). Hepatocellular carcinoma in women: probable lack of etiologic association with oral contraceptive steroids. Hepatology. (In the published literature, there were 34 reports of hepatocellular carcinoma [HCC] in women on OCCs, but relative risk is unknown; among 128 cases of HCC in women in files of Armed Forces Institute of Pathology between 1953 and 1980, 48 were below 40 years of age, of whom only 27% were on OCCs and 62% of these had fibrolamellar carcinoma, suggesting that the link between HCC with OCC use is due to chance).
Bühler H, Pirovino M, Akobiantz A, Altorfer J, Weitzel M, Maranta E, Schmid M. (1982). Regression of liver cell adenoma. A follow-up study of three consecutive patients after discontinuation of oral contraceptive use. Gastroenterology. (Found 4 cases of hepatic adenoma in young women between 1975-78, all on OCCs; one resected and three stopped OCCs and were followed, all regressed over 1-3 years).
Shar SR, Kew MC. (1982). Oral contraceptives and hepatocellular carcinoma. Cancer. (23 year old woman on OCCs for 22 months presented with acute rupture of hepatocellular carcinoma, no other risk factors, dying 2 years later of progressive cancer).
Kolb A. (1982). Benign liver tumors and oral contraceptives. Acta Chir Scand. (30 year old woman on OCCs for 15 years presented with abdominal mass found to be “orange” sized hepatic adenoma).
Freedman AN. (1982). Liver lesions and oral contraceptives. Can Med Assoc J. (32 year old woman presented with pain and multiple cavernous hemangiomas and a focal nodular hyperplasia with resolution after resection and stopping OCCs).
Zafrani ES, von Pinaudeau Y, Dhumeaux D. (1983). Drug-induced vascular lesions of the liver. Arch Intern Med. (Review of vascular lesions of liver associated with medications including OCCs: Budd Chiari syndrome, veno-occlusive disease, sinusoidal dilatation, peliosis hepatis, and vascular tumors).
Henderson BE, Preston-Martin S, Edmondson HA, Peters RL, Pike MC. (1983). Hepatocellular carcinoma and oral contraceptives. Br J Cancer. (Search for all deaths from liver cancer in women ages 18-39 in Los Angeles County from 1975-80 found 12 cases; 11 were interviewed and matched with controls; 3 were fibrolamellar; 1 occurred with adenoma and focal nodular hyperplasia; 10 cases had used OCCs and average duration was significantly longer than in controls[~5 vs ~2 years]).
Kerlin P, Davis GL, McGill DB, Weiland LH, Adson MA, Sheedy PF. (1983). Hepatic adenoma and focal nodular hyperplasia: clinical, pathologic, and radiologic features. Gastroenterology. (Retrospective analysis of 23 hepatic adenomas and 41 focal nodular hyperplasias (FNH) seen at the Mayo Clinic between 1961-80; 90% in women, mean age 34 years, OCC use in 80-83%; adenomas typically presented with pain and were larger [9 cm], FNH as an incidental finding and smaller [4 cm]; liver enzymes were usually normal; survival excellent; one woman with hepatic adenoma died 2 years later of hepatocellular carcinoma).
Lewis JH, Tice HL, Zimmerman HJ. (1983). Budd-Chiari syndrome associated with oral contraceptive steroids: review of treatment of 47 cases. Dig Dis Sci. (26 year old woman on OCCs for 7 year presented with 3 month history of fluid retention, edema and ascites which resolved clinically after stopping OCCs and use of aspirin and dipyridamole; review of literature and questionnaires sent to U.S. hepatologists identified 47 cases of Budd-Chiari syndrome associated with OCCs, some requiring surgical intervention: Case 4).
Forman D, Doll R, Peto R. (1983). Trends in mortality from carcinoma of the liver and the use of oral contraceptives. Br J Cancer. (Analyzed UK national death rates for liver tumors from 1958-81; liver tumors were rare, but there was a slight increase in rate among women ages 20 to 49 years between 1970 and 81; there were several possible explanations for this increase other than OCC use).
Gala KV, Griffin TW. (1983). Hepatomas in young women on oral contraceptives: report of two cases and review of the literature. J Surg Oncol. (Two cases: 40 year old woman with hepatocellular carcinoma [HCC] had taken OCCs for 8 years, stopping 3 years before presentation, successfully resected; 35 year old woman with metastatic HCC had been on OCCs for 12 years, died on chemotherapy; review of 25 cases in the literature).
Barrows GH, Christopherson WM. (1983). Human liver tumors in relation to steroidal usage. Environ Health Perspect. (Registry of liver tumors in young women since 1973 had 98 cases of focal nodular hyperplasia, 71 hepatic adenomas and 23 hepatocellular carcinomas; OCC use in >80% of all three groups).
Lieberman DA, Keefe LB, Stenzel P. (1984). Severe and prolonged oral contraceptive jaundice. J Clin Gastroenterol. (22 year old woman developed jaundice and pruritus after first cycle of OCCs with prolonged cholestatic course [bilirubin rising from ~7.0 to 19.5 mg/dL, ALT 180 to 291 U/L, Alk P ~170 to 556 U/L], requiring 6 months to resolve: Case 2).
Jacobs MB. (1984). Hepatic infarction related to oral contraceptive use. Arch Intern Med. (30 year old woman cigarette smoker on OCCs for 10 years developed abdominal pain, worsening ALT and Alk P, and was found to have hepatic artery thrombosis and liver infarcts, ultimately resolving after stopping OCCs).
Scragg RK, McMichael AJ, Seamark RF. (1984). Oral contraceptives, pregnancy and endogenous oestrogen in gall stone disease: a case-control study. Br Med J (Clin Res Ed). (Case controlled study of 200 hospitalized patients with gallstone disease; increased risk among young women who had taken OCCs, but decreased risk in older woman with a history of OCC use).
Scott LD, Katz AR, Duke JH, Cowan DF, Maklad NF. (1984). Oral contraceptives, pregnancy and focal nodular hyperplasia of the liver. JAMA. (36 year old woman on OCCs for 11 years developed hepatic mass which regressed on stopping OCCs, but arose again during a pregnancy; resection showed focal nodular hyperplasia with prominent central scar).
Schmitt FC, Luchsinger AE, Melo CR, Melo IS, Cechella MS. (1984). Arq Gastroenterol.
Mays ET, Christopherson W. (1984). Hepatic tumors induced by sex steroids. Semin Liver Dis. (Review of experience with 201 benign tumors of liver in women, ages 14 to 57; 98 were diagnosed as focal nodular hyperplasia, 2 adenoma and 23 hepatocellular carcinoma, 9 unclassified; history of OCC use in 82% regardless of histological diagnosis).
Jiménez Garrido MC, Aguinaga Manzanos MV, Miguel Velasco JE, Parada Herrero R, Placer Galan C, Sagredo Ruperez P, Soleto Saez E. (1984). Rev Esp Enferm Apar Dig. (52 year old woman on OCCs for 16 years presented with abdominal pain and laparotomy showed multiple adenomas).
Bretagne JF, Deugnier Y, Launois B, Gosselin M, Ferrand B, Gastard J. (1984). Gastroenterol Clin Biol. (31 year old on OCCs for 12 years developed hepatic mass that had features of focal nodular hyperplasia with areas of hepatocellular carcinoma with subsequent spread, rise in alpha-fetoprotein and death 9 months later).
Terpstra OT, ten Kate FJ, van Urk H. (1984). Long-term survival after resection of a hepatocellular carcinoma with lymph node metastasis and discontinuation of oral contraceptives. Am J Gastroenterol. (21 year old woman on OCCs for 2.5 years was found to have a 10 cm hepatocellular carcinoma that was resected; OCCs were stopped and she remained well during 6 years of follow-up despite the finding of a microscopic lymph node metastases).
Hromas RA, Srigley J, Murray JL. (1985). Clinical and pathological comparison of young adult women with hepatocellular carcinoma with and without exposure to oral contraceptives. Am J Gastroenterol. (Retrospective study of 29 young women with hepatocellular carcinoma seen between 1960-85 comparing those with [n=15] and without [n=14] estrogen exposure found minor differences, but suggested more benign course for those related to estrogens).
Eugene M, Chong MF, Genin R, Amat D. (1985). Mediterr Med. (29 year old woman presented with abdominal pain and bloating and was found to have ascites and varices; biopsy showed peliosis hepatis).
Spormann H, Willgeroth C, Tautenhahn P. (1985). Zentralbl Allg Pathol. (50 year old woman presented with hepatic rupture with massive peliosis and 8 cm tear; no mention of whether she was taking OCCs or estrogens).
Dean PJ, Haggitt RC, O’Hara CJ. (1985). Malignant epitheliod hemangioendothelioma of the liver in young women. Relationship to oral contraceptive use. Am J Surg Pathol. (Five cases of epitheliod hemangioendothelioma seen between 1980-83: all women usually presenting with right upper quadrant pain, all had taken OCCs for 4-7 years [up to 8 years before presentation], 3 died during follow up of disease progression).
Gonzalez F, Marks C. (1985). Hepatic tumors and oral contraceptives: surgical management. J Surg Oncol. (Retrospective analysis of 14 patients with benign liver tumors [88% adenomas]; 12 women, 11 on OCCs).
Flejou JF, Barge J, Menu Y, Degott C, Bismuth H, Potet F, Benhamou JP. (1985). Liver adenomatosis: an entity distinct from liver adenoma?. Gastroenterology. (Between 1979 and 1984, authors saw 5 patients with liver adenomatosis [3 men, 2 women not on OCCs] and 20 with adenoma [18 women, 14 on OCCs] suggesting a separate, possibly genetic, cause for adenomatosis).
Gordon SC, Reddy KR, Livingstone AS, Jeffers LJ, Schiff ER. (1986). Resolution of a contraceptive-steroid-induced hepatic adenoma with subsequent evolution into hepatocellular carcinoma. Ann Intern Med. (36 year old woman on OCCs for 14 years presented with 13 cm hepatic adenoma which decreased in size and became undetectable 2 years after stopping OCCs; 7 years later during cholecystectomy found to have a 4 cm mass with hepatocellular carcinoma, later metastasizing to peritoneum).
Neuberger J, Forman D, Doll R, Williams R. (1986). Oral contraceptives and hepatocellular carcinoma. Br Med J (Clin Res Ed). (Among 26 women less than 50 years old with hepatocellular carcinoma and with cirrhosis, 18 had used OCCs; compared to a control population relative risk for use of OCCs for more than 8 years was 4.4 in those with liver cancer; no increased risk with shorter durations of use).
Forman D, Vincent TJ, Doll R. (1986). Cancer of the liver and the use of oral contraceptives. Br Med J (Clin Res Ed). (Case control study of 30 women with liver cancer, 19 with hepatocellular carcinoma [HCC] and 11 with cholangiocarcinoma; relative risk for OCCs was 3.8 for HCC [increasing with greater years of use], but 0.3 for OCC use in cholangiocarcinoma).
Iverson O-E, Thoresen SØ. (1986). Oral contraceptives and hepatocellular carcinoma. Br Med J (Clin Res Ed). (Review of national records from Norway demonstrated rise in rates of hepatocellular carcinoma among women, but only in those >45 years, suggesting little effect of introduction of OCCs).
Brosens I, Johanisson E, Baulieu E-E, Benagiano G, Cooke ID, Goldzieher JW, Hammerstein J, et al. (1986). Oral contraceptives and hepatocellular carcinoma. Br Med J (Clin Res Ed). (International Committee for Research in Reproduction comments that studies of Neuberger and Forman still show that hepatocellular carcinoma is very rare and the association with OCCs still unproven).
Valla D, Le MG, Poynard T, Zucman N, Rueff B, Benhamou JP. (1986). Risk of hepatic vein thrombosis in relation to the recent use of oral contraceptives: a case control study. Gastroenterology. (Case control study of 33 cases of hepatic vein thrombosis and 128 matched controls identified via questionnaires to 25 French Hepatology centers; OCC use in 54% of cases, 31% of controls for odds ratio of 2.37; 72% of OCC related cases had another underlying predisposing condition).
Grigsby P, Meyer JS, Sicard GA, Huggins MB, Lamar DJ, DeSchryver-Kecskemeti K. (1987). Hepatic adenoma within a spindle cell carcinoma in a woman with a long history of oral contraceptives. J Surg Oncol. (38 year old on OCCs for 8 years presented with a hepatic mass found to be hepatic adenoma within a multicentric anaplastic spindle cell tumor).
Kreitner KF, Thelen M, Schild H, Heintz A, Störkel S. (1987). Dtsch Med Wochenschr. (Review of literature and 19 local cases of focal nodular hyperplasia; found 886 cases, mostly published in previous 15 years, 82% women, mean age 32 years, 58% on OCCs; 0.3 to 24 cm [mean=6 cm], 35% with symptoms, 20% with palpable mass, prognosis good, rare reports of subsequent malignancy).
Ishak KG, Zimmerman HJ. (1987). Hepatotoxic effects of the anabolic/androgenic steroids. Semin Liver Dis. (Extensive review of hepatotoxicity of androgenic steroids).
van Erpecum KJ, Janssens AR, Kreuning J, Ruiter DJ, Kroon HM, Grond AJ. (1988). Generalized peliosis hepatis and cirrhosis after long-term use of oral contraceptives. Am J Gastroenterol. (43 year old woman with epigastric discomfort and fatigue on OCCs for 12 years had a large liver and abnormal liver scan, [bilirubin 1.0 mg/dL, ALT 21 U/L, Alk P 376 U/L], liver biopsy showing peliosis; OCCs were stopped, but she developed progressive liver disease with high Alk P [1208 U/L] but minimal ALT elevations [45 U/L], ultimately requiring liver transplantation 11 years later).
Heresbach D, Deugnier Y, Brissot P, Bourel M. (1988). Ann Gastroenterol Hepatol (Paris). (23 year old woman on OCCs for 7 years was admitted for abdominal pain [ALT 149 U/L, Alk P 37 U/L, bilirubin not provided] and liver biopsy showed sinusoidal dilatation without inflammation, necrosis or fibrosis], symptoms and ALT elevations resolving within 8 days of stopping OCCs).
Marks WH, Thompson N, Appleman H. (1988). Failure of hepatic adenomas (HCA) to regress after discontinuance of oral contraceptives. An association with focal nodular hyperplasia (FNH) and uterine leiomyoma. Ann Surg. (Three cases; 34 to 37 year old women on OCCs for 2-3 years [but 6-10 years before clinical presentation] found to have hepatic adenomas, two also had focal nodular hyperplasia).
Valla D, Benhamou JP. (1988). Liver diseases related to oral contraceptives. Dig Dis. (Review of hepatic complications of OCCs including intrahepatic cholestasis, adenoma, focal nodular hyperplasia, hepatocellular carcinoma, sinusoidal dilatation, Budd Chiari syndrome and portal vein thrombosis).
Ferrara BE, Rutland ED. (1988). Liver tumor in long-term user of oral contraceptives. Postgrad Med. (36 year old woman on OCCs for 6 years presented with rupture of 15 x10 cm hepatic adenoma).
Conter RL, Longmire WP. (1988). Recurrent hepatic haemangiomas: possible association with estrogen therapy. Ann Surg. (4 cases of recurrent giant hepatic hemangiomas [>4 cm]; 3 in women; each with recurrence many years later while on chronic estrogen therapy).
Balázs M. (1988). Sinusoidal dilatation of the liver in patients on oral contraceptives. Electron microscopic study of 14 cases. Exp Pathol. (Electron microscopic analysis of 14 liver biopsies from 37 women on OCCs for 2-12 years undergoing routine cholecystectomy who were found to have hepatomegaly; enlarged but intact endothelial cells, slight collagen, hepatocytes normal, sinusoids empty and capillarized).
Palmer JR, Rosenberg L, Kaufmann DW, Warshauer NE, Stolley P, Shapiro S. (1989). Oral contraceptive use and liver cancer. Am J Epidemiol. (Among 9 cases of hepatocellular carcinoma in women 19 to 54 years old who were identified between 1977-85 in five US medical centers, 89% were on OCCs compared to 36% of controls, for relative risk of 20).
Foitl DR, Hyman G, Lefkowitch JH. (1989). Jaundice and intrahepatic cholestasis following high-dose megestrol acetate for breast cancer. Cancer. (Woman with breast cancer treated with high doses of megestrol [progesterone] developed abnormal liver tests [ALT 160 U/L, Alk P 324 U/L] five weeks later, followed by jaundice [bilirubin rising to 16 mg/dL], dying suddenly a few days later and having multiple metastases in liver).
Gyorffy EJ, Bredfeldt JE, Black WC. (1989). Transformation of hepatic cell adenoma to hepatocellular carcinoma due to oral contraceptive use. Ann Intern Med. (58 year old on OCCs for 19 years found to have 8 by 12 cm adenoma; stopped OCCs, but 2-3 years later had rising alpha-fetoprotein and biopsy showed hepatocellular carcinoma).
La Vecchia C, Negri E, Parazzini F. (1989). Oral contraceptives and primary liver cancer. Br J Cancer. (Case control study from Italy identified 21 women [ages 32 to 59 years] with liver cancer diagnosed between 1984-87; only 4 cases [19%] used OCCs compared to 8% of controls; relative risk for OCC use <5 years was 1.8 and for >5 years 8.3; but based on few cases).
(1989). Combined oral contraceptives and liver cancer. The WHO Collaborative Study of Neoplasia and Steroid Contraceptives. Int J Cancer. (Results of hospital based, case control study of 122 cases of primary liver cancer and 802 matched controls; no increase in risk associated with OCC use, but most cases were from areas of the world with high rates of hepatitis B and most OCC use was for a short duration).
Kew MC, Song E, Mohammed A, Hodkinson J. (1990). Contraceptive steroids as a risk factor for hepatocellular carcinoma: a case/control study in South African black women. Hepatology. (Case control study in 46 women, ages 19 to 54 years with hepatocellular carcinoma from an endemic area for hepatitis B; 32% of cases and 37% of controls had used OCCs, whereas 41% of cases versus 9% of controls had HBsAg in serum).
Korula J, Yellin A, Knel G, Camporiofi G, Nichols P. (1991). Hepatocellular carcinoma coexisting with hepatic adenoma–Incidental discovery after long-term oral contraceptive use. West J Med. (40 year old woman on OCCs for 15 years and estrogens for 6 years found to have an incidental hepatic mass, which on resection was adenoma with areas of hepatocellular carcinoma).
Prentice RL. (1991). Epidemiologic data on exogenous hormones and hepatocellular carcinoma and selected other cancers. Prev Med. (Review of epidemiologic evidence linking OCCs and exogenous estrogen use to cancers: combing 4 case control studies of hepatocellular carcinoma found relative risk of 2.6 for ever using OCCs, 9.6 for prolonged use).
Adam G, Lesser T, Neumann R. (1991). Zentralbl Chir. (44 year old woman on OCCs for 13 years developed abdominal pain and anemia leading to diagnosis of hepatic bleeding from peliosis hepatis, with fatal outcome after attempted resection).
Tao LC. (1992). Are oral contraceptive-associated liver cell adenomas premalignant?. Acta Cytol. (Among 1670 patients undergoing fine needle aspiration of diagnosis of liver masses between 1977-90 in Toronto, 99 patients had hepatocellular carcinoma [3 on OCCs] and 9 had hepatic adenoma [all on OCCs]).
Wedén M, Glaumann H, Einarsson K. (1992). Protracted cholestasis probably induced by oral contraceptive. J Intern Med. (35 year old woman on OCCs for 14 years found to have elevations in Alk P 4 times ULN, but normal bilirubin and ALT; Alk P improved after stopping, but was still elevated 10 years later).
Stanford JL, Thomas DB. (1992). The WHO Collaborative Study of Neoplasia and Steroid Contraceptives. Reproductive factors in the etiology of hepatocellular carcinoma. Cancer Causes and Control. (Results from hospital based case control study in 4 developing countries of 83 patients with hepatocellular carcinoma [HCC] vs 596 controls found having multiple full term pregnancies, but not use of OCCs was associated with HCC).
Hsing AW, Hoover RN, McLaughlin JK. (1992). CoChien HT, Wacholder S, Blot W, Fraumeni JF Jrl. Oral contraceptives and primary liver cancer among young women. Cancer Causes Control. (Analysis of National Mortality Followback Survey, identifying 76 cases of primary liver cancer, 22 bile duct cancers and 629 controls; OCC use in 54% of cases vs 44% of controls, odds ratio of 1.6 for ever use and 2.0 for >10 years of use).
Le Bail B, Jouhanole H, Deugnier Y, Salame G, Pellegrin JL, Saric J, Balabaud C, Bioulac Sage P. (1992). Liver adenomatosis with granulomas in two patients on long-term oral contraceptives. Am J Surg Pathol. (Two cases of hepatic adenomatosis in women, 39 and 52 years old, on OCCs for 12 and 18 years; one continued to have new lesions during follow up off of OCCs).
Tavani A, Negri E, Parazzini F, Franceschi S, La Vecchia C. (1993). Female hormone utilization and risk of hepatocellular carcinoma. Br J Cancer. (Case control study of 82 Italian women [ages 28 to 73 years] with diagnosis of hepatocellular carcinoma; relative risk was OCC users was 2.6 and risk increased with duration of use, but overall use was low [21%]).
Thijs C, Leffers P, Knipschild P. (1993). Oral contraceptive use and the occurrence of gallstone disease–a case-control study. Prev Med. (Case control study of gallstone disease from the Netherlands matched 110 cases with 355 controls for OCC use and duration; after adjusting for many confounders, found a mild early effect of OCC [first 5 years] use that disappeared with time).
Thijs C, Leffers P, Knipschild P. (1993). Oral contraceptives and the risk of gallbladder disease: a meta-analysis. Am J Public Health. (Metaanalysis identified 25 studies of association of OCC use and gallstone disease; many inconsistencies in conclusions and many confounding factors including latency from development of gallstones and appearance of symptoms and changes in OCC formulations; concluded that OCC use probably had a weak effect, if any at all).
Ferrell LD. (1993). Hepatocellular carcinoma arising in a focus of multilobular adenoma. A case report. Am J Surg Pathol. (29 year old woman with abdominal pain, hepatic mass and Alk P >2000 U/L, found to have an 18 cm hepatic adenoma within which was a 5 cm hepatocellular carcinoma; patients was without evidence of recurrence 4 years later).
Reyes H, Simon FR. (1993). Intrahepatic cholestasis of pregnancy: an estrogen-related disease. Semin Liver Dis. (Review of clinical features, epidemiology, pathogenesis and management of intrahepatic cholestasis of pregnancy and its relation to OCCs and estrogens, including effects of ursodiol in improving pruritus, and ALT and bile salt levels).
Lindgren A, Olsson R. (1993). Liver damage from low-dose oral contraceptives. J Intern Med. (Analysis of adverse drug reaction reports to Swedish Registry for 1965-75 showed marked decrease in reports of liver injury from OCCs during period of lowering estrogen dose in pill; fell to 1 per million OCC cycles).
Chu G, Farrell GC. (1993). Portal vein thrombosis associated with prolonged ingestion of oral contraceptive steroids. J Gastroenterol Hepatol. (38 year old woman smoker on OCCs for 24 years developed portal vein thrombosis, responding to anticoagulation and stopping OCCs).
Grodstein F, Colditz GA, Hunter DJ, Manson JE, Willett WC, Strampfer MJ. (1994). A prospective study of symptomatic gallstones in women: relation with oral contraceptives and other risk factors. Obstet Gynecol. (Analysis of Nurses Health Study cohort based upon questionnaires found 425 cases of symptomatic gallstones, showed minimal association with long term OCC use [relative risk 1.5], but strong association with higher body mass index and weight gain; lesser association with smoking and parity).
Rabe T, Feldmann K, Grunwald K, Runnebaum B. (1994). Liver tumors in women on oral contraceptives. Lancet. (Since 1971, 637 cases of liver tumors in women on OCCs, but no cases reported with use of cyproterone).
Herman P, Machado MA, Volpe P, et al. (1994). Rev Hosp Clin Fac Med Sao Paulo. (Two cases of hepatic adenoma with focal areas of hepatocellular carcinoma in 30 and 37 year old women on OCCs for 15 and 20 years).
Gisbert PJ, González A, Moreira V, Sanromán LA, Hernández F, Cano A. (1994). Rev Esp Enferm Dig. (40 year old woman on OCCs for 3 years presented with abdominal pain found to have spontaneous hepatic hematomas due to widespread peliosis).
Colditz GA. (1994). Oral contraceptive use and mortality during 12 years of follow-up: the Nurses’ Health Study. Ann Intern Med. (Analysis of Nurse’s Health Study: in 166,755 women found no increase in risk of mortality associated with OCC even after multivariable adjustment).
Mant JWF, Vessey MP. (1995). Trends in mortality from primary liver cancer in England and Wales 1975-92: influence of oral contraceptives. Br J Cancer. (Age specific mortality trends for primary liver cancer in women remained constant in England and Wales between 1975 and 1992 in all age groups; death rates being ~1.4 per million in women 25 to 34 years old).
Staub PG, Leibowitz CB. (1996). Peliosis hepatis associated with oral contraceptive use. Australas Radiol. (35 year old on OCCs for several years developed abdominal pain with multiple liver lesions on ultrasound and CT, biopsy showing peliosis, improvement but not resolution on ultrasound 6 months later; no liver test results provided).
Perret AG, Mosnier JF, Porcheron J, Cuilleron M, Berthoux P, Boucheron S, Audigier JC. (1996). Role of oral contraceptives in the growth of a multilobular adenoma associated with a hepatocellular carcinoma in a young woman. J Hepatol. (24 year old woman on OCCs for 3 years presented with abdominal pain and found to have a 14 cm adenoma with focal HCC which was resected).
Waetjen LE, Grimes DA. (1996). Oral contraceptives and primary liver cancer: temporal trends in three countries. Obstet Gynecol. (Analysis of primary liver cancer deaths from US, Japan and Sweden with several hundred million woman-years of exposures to OCCs found no support for role of OCCs in causing hepatocellular carcinoma).
Fiel MI, Min A, Gerber MA, Faire B, Schwartz M, Thung SN. (1996). Hepatocellular carcinoma in long-term oral contraceptive use. Liver. (4 women on OCCs for 8-15 years presented with hepatocellular carcinoma with accompanying cirrhosis; two died and two survived long term after resection and stopping OCCs).
Persson I, Yuen J, Bergkivist L, Schairer C. (1996). Cancer incidence and mortality in women receiving estrogen-replacement therapy—long-term follow-up of a Swedish cohort. Int J Cancer. (Among 22,579 women on estrogen replacement therapy followed for an average of 13.2 years, 2330 cancers occurred, including 14 liver cancers, lower incident rate ratio [0.6] than expected).
Benhamou JP. (1997). Gastroenterol Clin Biol. (Review of the literature on the association of hepatic adenoma, focal nodular hyperplasia and hepatic angioma with use of birth control pills, with recommendations on management).
Hannaford PC, Kay CR, Vessey MP, Painter R, Mant J. (1997). Combined oral contraceptives and liver disease. Contraception. (Analysis of two large prospective studies of OCC use from the UK [>200,000 women-years] found low rate of liver disease and no association with OCC use; in one study, a possible increased risk for mild liver disease during first 4 years of use).
The Collaborative MILTS Project Team. (1997). Oral contraceptives and liver cancer. Results of the Multicentre International Liver Tumor Study (MILTS). Contraception. (Case control study among 317 women <65 years old with hepatocellular carcinoma; relative risk among OCC users was 0.75 compared to controls with no increase with longer use; important risk factors were hepatitis B and C; however, after excluding these risk factors, the relative risk was increased for women who used OCCs for >6 years).
Heinemann LA, Weimann A, Gerken G, Thiel C, Schlaud M, DoMinh T. (1998). Modern oral contraceptive use and benign liver tumors: the German Benign Liver Tumor Case-Control Study. Eur J Contracept Reprod Health Care. (51 hepatic adenomas and 143 focal nodular hyperplasias [FNHs] accrued by 15 medical centers in Germany between 1990-97 and compared to 240 controls; OCC use reported in 94% of adenoma and 96% of FNH cases compared to 70% of controls, but odds ratios were not significant after controlling for age; slight increase in FNH with longer duration of use).
Meunier F, Boyer L, Abergel A, Perez N, Ravel A, Lhopital F, Viallet JF. (1998). J Radiol. (47 year old woman on OCCs for 7 years found to have 5 cm focal nodular hyperplasia, which persisted for 2 years and then regressed on stopping OCCs and was no longer radiologically evident 5 years later).
Meissner K. (1998). Hemorrhage caused by ruptured liver cell adenoma following long-term oral contraceptives: a case report. Hepatogastroenterology. (41 year old woman on OCCs for 14 years presented with ruptured hepatic adenoma requiring emergency resection).
Dourakis SP, Tolis G. (1998). Sex hormonal preparations and the liver. Eur J Contracept Reprod Health Care. (Review of sex hormones and liver injury; estrogen complications include cholestasis, cholelithiasis, Budd-Chiari syndrome, peliosis, adenomas, focal nodular hyperplasia and HCC).
Ye MQ, Suriawinata A, Ben Haim M, Parsons R, Schwartz ME. A. (1999). 42-year-old woman with liver masses and long-term use of oral contraceptives. Semin Liver Dis. (42 year old woman on OCs for 25 years presented with an abdominal mass which on surgery was found to be 2 adenomas with focal areas of hepatocellular carcinoma, successfully resected).
Naduka CC. (1999). Hepatic adenoma following short period of oral contraceptive use. J Am Board Fam Pract.
Makhlouf HR, Ishak KG, Goodman ZD. (1999). Epithelioid hemangioendothelioma of the liver: a clinicopathologic study of 137 cases. Cancer. (Analysis of 137 cases of epithelioid hemangioendothelioma from the Armed Forces Institute of Pathology; mean age 47 years, 61% women; incidental finding in 42%, symptoms if present usually pain, ~50% 5-year survival, little information on OCCs, but unlikely to be important).
De Block CEM, De Leeuw IV, Van Gaal LF. (1999). Premenstrual attacks of acute intermittent porphyria: hormonal and metabolic aspects–a case report. Eur J Endocrinol. (38 year old woman with acute intermittent porphyria had several premenstrual attacks resolving with luteinizing hormone-releasing hormone analogue therapy [triptorelin]).
Follmann M, Heinemann LA, Bauerfeind A, Garbe E. (2000). Treatment with potentially hepatotoxic drugs and the risk of hepatocellular carcinoma: results of a European case-control study. Pharmacoepidemiol Drug Saf. (Further analysis of the international case control study of 317 cases of hepatocellular carcinoma and 1060 controls [MILTS], found no association or increase risk of the cancer with common medication use: nitrofurantoin, antidiabetic medications, methyldopa, clofibrate or immunosuppressive agents).
Minnema MC, Janssen HL, Niermeijer P, de Man RA. (2000). Budd-Chiari syndrome: combination of genetic defects and the use of oral contraceptives leading to hypercoagulability. J Hepatol. (18 year old woman on OCCs for 3 years developed abdominal discomfort and swelling diagnosed as hepatic vein thrombosis and was found to be heterozygous for Factor V Leiden and for Factor II G20210A mutation).
Mathieu D, Kobeiter H, Maison P, Rahmouni A, Cherqui D, Zafrani ES, Dhumeaux D. (2000). Oral contraceptive use and focal nodular hyperplasia of the liver. Gastroenterology. (Analysis of 216 women with focal nodular hyperplasia seen between 1989 and 1998; neither size nor number of masses were associated with OCC use, and neither continued use or pregnancy were associated with tumor).
Siepmann M, Kirch W. (2000). Dtsch Med Wochenschr. (51 year old woman developed generalized pruritus while on estrogen-progesterone hormonal replacement therapy for 7 years with normal ALT, Alk P and bilirubin [0.4 mg/dL], unresponsive to antihistamines and steroid creams, resolving rapidly with stopping hormone therapy).
Westhoff C, Britton JA, Gammon MD, Wright T, Kelsey JL. (2000). Oral contraceptive and benign ovarian tumors. Am J Epidemiol. (In a case control study from 6 New York medical centers, OCC use was associated with a decreased risk of developing benign ovarian tumors).
Tajada M, Nerín J, Ruiz MM, Sánchez-Dehesa M, Fabre E. (2001). Liver adenoma and focal nodular hyperplasia associated with oral contraceptives. Eur J Contracept Reprod Health Care. (40 year old woman on OCCs for 15 years found to have 8 cm liver mass on incidental ultrasound; stopping OCCs resulted in no change in size and surgery revealed focal nodular hyperplasia).
Wang SY, Ruggles S, Vade A, Newman BM, Borge MA. (2001). Hepatic rupture caused by peliosis hepatis. J Pediatr Surg. (3 year old boy with “myotubular myopathy” developed abdominal distension and shock; found to have ruptured hepatic mass, believed to be peliosis hepatis; recovered with surgical and radiologic intervention).
Aseni P, Sansalone CV, Sammartino C, Di Benedetto F, Carrafiello G, Giacomoni A, Osio C, et al. (2001). Rapid disappearance of hepatic adenoma after contraceptive withdrawal. J Clin Gastroenterol. (25 year old woman on OCCs for 8 years found to have abnormal Alk P and GGT; ultrasound showed 5 cm mass that disappeared 9 months after stopping OCCs).
D'Souza RE, Guillebaud J. (2002). Risks and benefits of oral contraceptive pills. Best Pract Res Clin Obstet Gynaecol. (Review of risks of OCCs including venous thromboembolism, coronary and cerebrovascular disease and hypertension; breast cancer, liver tumors [3/100,00 users per year], hepatocellular carcinoma [uncertain association] and jaundice [1,10,000 users] but these risks may be lower with current, low dose pills).
Scalori A, Tavanni A, Gallus S, La Vecchia C, Colombo M. (2002). Oral contraceptives and the risk of focal nodular hyperplasia of the liver: a case-control study. Am J Obstet Gynecol. (Case control study of 23 Italian women with focal nodular hyperplasia; 83% of cases and 59% controls reported OCC use; odds ratio was 2.5, and 4.5 for >3 years of use).
Andersson C, Innala E, Backstrom T. (2003). Acute intermittent porphyria in women: clinical expression, use and experience of exogenous sex hormones. A population-based study in northern Sweden. J Intern Med. (Female sex hormones appear to increase porphyrin precursors and may precipitate attacks of acute intermittent porphyria [AIP]; questionnaires completed by 166 women with AIP in Sweden; 91 had symptomatic disease; mean age of onset 25 years and reduction in symptoms after menopause in 50%; pregnancy appeared to have little effect and only 25% reported precipitation of attacks with OCCs; hormonal replacement therapy had no effect).
Ito M, Sasaki M, Wen CY, Nakashima M, Ueki T, Ishibashi H, Yano M, et al. (2003). Liver cell adenoma with malignant transformation: a case report. World J Gastroenterol. (57 year old found to have adenoma with area of hepatocellular carcinoma; only OCC use was for one month 27 years previously).
Mansvelt B, Etienne PY, Bertrand C, Henrion J, Gerard R. (2003). Hepatocellular carcinoma associated with precocious puberty and oral contraceptives. A case report. Acta Chir Belg. (36 year old woman on OCCs for 18 years presented with sudden onset of abdominal pain and was found to have well differentiated hepatocellular carcinoma in a liver without fibrosis; resected and was alive without recurrence 4 years later).
Gemer O, Moscovici O, Ben-Horin CL, et al. (2004). Oral contraceptives and liver hemangioma: a case-control study. Acta Obstet Gynecol Scand. (Case control study of 40 women with liver hemangiomas and 109 controls; OCC use in 30% vs 27%).
Hung NR, Chantrain L, Dechambre S. (2004). Peliosis hepatis revealed by biliary colic in a patient with oral contraceptive use. Acta Chir Belg. (42 year old woman on OCCs for several years developed right upper quadrant pain and tenderness with normal liver tests and multiple cysts and lesions on ultrasound and magnetic resonance [possible peliosis hepatis], decreasing after stopping OCCs).
Yu MC, Yuan JM. (2004). Environmental factors and risk for hepatocellular carcinoma. Gastroenterology. (Review of risk factors for hepatocellular carcinoma; highest risk with hepatitis B and C [odds ratios 20-24], but also aflatoxin exposure and alcohol use; 8 case control studies in young, non-cirrhotic women for role of OCCs, summary odds ratio of 2.5 for ever using OCCs and 5.8 for longest duration of use; this effect is hard to show in high endemic areas).
Gomes MP, Deitcher SR. (2004). Risk of venous thromboembolic disease associated with hormonal contraceptives and hormone replacement therapy: a clinical review. Arch Intern Med. (Systematic review of risk of thromboembolic disease with oral contraceptive use; risk of venous thromboses appears to be increased during the first 6-12 months of therapy, is higher in older women, is higher with higher doses of estrogens, in patients with inherited hypercoagulable states [99 fold with factor V Leiden and 16-fold with the prothrombin G20210A mutation]; similar increase in risk [~2.1] was also found for hormonal replacement therapy in the Women’s Health Initiative).
Zucman-Rossi J. (2004). Genetic alterations in hepatocellular adenomas: recent findings and new challenges. J Hepatol. (Review of role of HNF1α mutations in adenomatosis; high rate of double, inactivating, somatic mutations in HNF1α in adenomas linked to birth control pills).
Hashimoto L, Dabbs A, Sewell P, Doherty M. (2004). Resection and radiofrequency ablation of multiple liver adenomas secondary to anti-conceptive pills. Hepatogastroenterology. (25 year old woman on OCCs presented with multiple hepatic adenomas, some resected and some treated with radiofrequency ablation).
Anand V, Gorard DA. (2005). Norethisterone-induced cholestasis. QJM. (Two cases of cholestatic liver injury in women receiving progesterone contraceptive only; 18 and 34 year old woman with onset of jaundice 2 weeks and 4 years after starting norethisterone [initial bilirubin 2.5 and 1.9 mg/L, ALT 540 and AST 179, Alk P 102 and 532 U/L], resolving within 2-4 months of stopping).
Lam CM, Yong JL, Chan AO, Ng KK, Poon RT, Liu CL, Lo CM, et al. (2005). Better survival in female patients with hepatocellular carcinoma: oral contraceptive pills related?. J Clin Gastroenterol. (In multivariate analysis of determinants of survival among 3,171 patients with hepatocellular carcinoma, female sex, fewer tumor nodules, smaller size, no vascular or other organ invasion and lack rupture were associated with survival).
Cirillo DJ, Wallace RB, Rodabough RJ, Greenland P, LaCroix AZ, Limacher MC, Larson JC. (2005). Effect of estrogen therapy on gallbladder disease. JAMA. (Analysis of Women’s Health Initiative postmenopausal hormone trial; among 22,579 women, higher rate of gallbladder events in women who received estrogens, separating after one year with hazard ratio of 1.8; progesterone did not appear to increase the rate further).
Maréchal R, Taccone FS, Bourgeois N, Hittelet A. (2005). Rev Med Brux.
Ruiz López D, Sánchez Salvador J, Fernández Martín C, Antón Díaz E. (2005). Aten Primaria.
Giannitrapani L, Soresi M, La Spada E, Cervello M, D'Alessandro N, Montalto G. (2006). Sex hormones and risk of liver tumor. Ann N Y Acad Sci. (Review of relationship of androgen and estrogen use and liver tumors. Hemangiomas occur more commonly in women [5:1] as does focal nodular hyperplasia [8:1] but their link to estrogens is controversial; adenomas are clearly linked to estrogen use and are rare in men; hepatocellular carcinoma is more common in men than women [9:1 in some studies] and estrogens appear to increase the risk slightly with an odds ratio of 2.5 for any use and 5.8 for long term use).
La Vecchia C, Tavani A. (2006). Female hormones and benign liver tumours. Dig Liver Dis. (Review of literature linking estrogen use and hepatic adenomas, focal nodular hyperplasia and hemangiomas).
Maheshwari S, Sarraj A, Kramer J, El-Serag HB. (2007). Oral contraception and the risk of hepatocellular carcinoma. J Hepatol. (Metaanalysis of studies on OCCs and hepatocellular carcinoma; 12 case control studies, pooled estimate of odds ratio of 1.57, but overall the evidence “is inconclusive”).
Gutiérrez Santiago M, García Ibarbia C, Nan DN, Hernández JL. (2007). Rev Clin Esp. (45 year old woman on OCCs for 9 years found to have multiple lesions in the liver due to peliosis, with partial resolution on stopping OCCs).
Dunn JM, McNair A. (2007). Prolonged cholestasis following successful removal of common bile duct stones: beware patients on estrogen therapy. World J Gastroenterol. (Two women with prolonged cholestasis after successful removal of common duct stones by ERCP, perhaps exacerbated by OCCs or hormonal replacement therapy).
Proctor DD, Henderson KJ, Dziura JD, White RI. (2008). Hormonal therapy for the treatment of gastrointestinal bleeding in hereditary hemorrhagic telangiectasia. J Clin Gastroenterol. (Case report of 51 year old woman with hereditary hemorrhagic telangiectasia [HHT] requiring multiple blood transfusions and iron because of gastrointestinal bleeding, had marked decrease in transfusion requirements within 4 months of starting OCCs).
Hay JE. (2008). Liver disease in pregnancy. Hepatology. (Review of pregnancy related liver disease including intrahepatic cholestasis of pregnancy defined by pruritus and elevated bile acid levels arising in second half of pregnancy, 25% with jaundice, resolving with delivery, typically recurring with subsequent pregnancies; 15% of cases linked to ABC B4 mutations; treatment includes ursodiol).
Bioulac-Sage P, Laumonier H, Laurent C, Zucman-Rossi J, Balabaud C. (2008). Hepatocellular adenoma: what is new in 2008. Hepatol Int. (Several gene mutations have been associated with hepatic adenomas some of which have distinct clinical phenotypes; [1] mutations in hepatocyte nuclear factor [HNF] 1α are found in 35% of adenomas, usually with steatosis and little inflammation; [2] β catenin gene mutations occur in 10% of adenomas and are associated with cytological abnormalities, without steatosis and with a higher rate of malignant transformation; [3] inflammatory adenomas are associated with increases in C-reactive protein in 40-50% of cases; [4] others, ~10% of cases; germline HNF1α mutations are associated with multiple liver adenomatosis and early onset type 2 diabetes [MODY3]).
Perarnau JM, Bacq Y. (2008). Hepatic vascular involvement related to pregnancy, oral contraceptives, and estrogen replacement therapy. Semin Liver Dis. (Review of vascular diseases of the liver and role of pregnancy, oral contraceptives and hormonal replacement therapy).
Meier Y, Zodan T, Lang C, Zimmermann R, Kulla K, Ublick GA, Meier PJ, et al. (2008). Increased susceptibility for intrahepatic cholestasis of pregnancy and contraceptive-induced cholestasis in carriers of the 1331T>C polymorphism in the bile salt export pump. World J Gastroenterol. (21 women with pregnancy- and 4 with OCC-associated cholestasis were assessed for variants in BSEP [ABC B11], MDR3 [ABC B4] and MRP2 [ABC C2]; no specific mutations were found in ABC C2 or B4, but all OCC related cases were homozygous for a single polymorphism in ABC B11, vs 57% of pregnancy-associated and 20% of controls).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 cases were attributed to an estrogen containing preparation).
Kapp N, Tilley IB, Curtis KM. (2009). The effects of hormonal contraceptive use among women with viral hepatitis or cirrhosis of the liver: a systematic review. Contraception. (Scant data are available, but most suggests that OCCs have little effect on the course and outcome of either acute or chronic viral hepatitis).
Bacq Y, Gendrot C, Perrotin F, Lefrou L, Chretien S, Vie-Buret V, Brechot MC, et al. (2009). ABCB4 gene mutations and single-nucleotide polymorphisms in women with intrahepatic cholestasis of pregnancy. J Med Genet. (Analysis of ABC B4 [flippase: MDR3] sequences in 50 women with intrahepatic cholestasis of pregnancy; 16% had gene mutations, but no distinguishing clinical features between those with and without ABC B4 mutations).
Geenes V, Williamson C. (2009). Intrahepatic cholestasis of pregnancy. World J Gastroenterol. (Intrahepatic cholestasis of pregnancy occurs worldwide [~1% of pregnancies], but is most common in Chile [1.5-4%] and Scandinavia; higher rates in twin pregnancies and in winter months, and familial associations with gallstones; arises usually in third trimester and resolves within 2 days of delivery; jaundice in 10-15% but rarely severe; ALT elevated 2-10 fold but not always; Alk P is elevated in normal pregnancy; bile acids invariably elevated; genomic studies suggest enormous heterogeneity; proportion linked to ABC B4 and ABC B11).
Rebouissou S, Amessou M, Couchy G, Poussin K, Imbeaud S, Pilati C, Izard T, Balabaud C, Bioulac-Sage P, Zucman-Rossi J. (2009). Frequent in-frame somatic deletions activate gp130 in inflammatory hepatocellular tumours. Nature. (A subset of hepatic adenomas have an inflammatory phenotype and were found to have elevations in acute phase reactants which led to identification of somatic deletions in gp130, a receptor in the IL6 signaling pathway and mutations activated STAT3 and downstream acute phase inflammatory genes).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, ethinylestradiol with levonorgestrel accounted for 43 cases [ranking 27th], with an adjusted odds ratio of 1.9 compared to controls).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, 1 case was attributed to an OCC).
Elouni B, Ben Salem C, Zamy M, Ganne N, Beaugrand M, Bouraoui K, Biour M. (2010). Cytolytic hepatitis possibly related to levonorgestrel/ethinylestradiol oral contraceptive use: 2 case reports. Ann Pharmacother. (Two women, ages 28 and 29, developed marked ALT elevations with no jaundice or Alk P elevations 11 and 8 months after starting OCCs, ALT levels increasing [from 7 to 31 times ULN and from 2 to 23 times ULN] as long as OCCs were continued and resolving within 3-4 weeks once stopped).
Tornai I. (2010). Orv Hetil. (Review of risk factors for hepatocellular carcinoma mentions that OCCs may play a role in some cases).
Jaffar R, Pechet L, Whalen GF, Banner BF. (2010). Spontaneous hepatic hemorrhage secondary to prolonged use of oral contraceptives. Pathol Res Pract. (45 year old woman who had taken OCCs for 18 years suffered a spontaneous subcapsular hematoma not related to tumor, peliosis or known trauma).
Pauli-Magnus C, Meier PJ, Stieger B. (2010). Genetic determinants of drug-induced cholestasis and intrahepatic cholestasis of pregnancy. Semin Liver Dis. (Review of pathogenesis of cholestatic liver disorders including intrahepatic cholestasis of pregnancy, which has been linked to genetic variants in the bile salt exporter protein [BSEP, ABC B11]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to estrogens or OCCs).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino RA, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Summary of 176 published cases of drug induced liver injury from 9 South American countries implicated a total of 53 drugs, 4 cases being due to estrogens, progestins or birth control pills, all of which were from Chile).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 [0.7%] were attributed to estrogens or OCCs, all female, ages 16 to 55 years [median 22], onset after 13-70 days [median 27], bilirubin 0.7-12.4 mg/dL, ALT 66-520 U/L, Alk P 54-241, 5 with itching, 3 with jaundice, mild-to-moderate in severity, resolving in all, 4 highly likely and 2 probable).
Loulergue P, Coriat R, Mir O. (2015). Recurrent transaminitis induced by oral contraceptives during HIV infection. Ann Pharmacother. (45 year old HIV positive woman on long term antiretroviral therapy developed abnormal liver tests without symptoms one month after starting oral contraceptives of ethinyl estradiol and levonorgestrel [bilirubin normal, ALT 17 times ULN], resolving within 3 weeks of stopping and then recurring several years later within 2 weeks of restarting ethinyl estradiol with norgestrel [ALT 12 times ULN], again resolving rapidly upon stopping).
Bourgeois AL, Auriche P, Palmaro A, Montastruc JL, Bagheri H. (2016). Risk of hormonotherapy in transgender people: Literature review and data from the French Database of Pharmacovigilance. Ann Endocrinol (Paris). (Review of the literature and adverse event registries on medical regimens for transgender individuals, trans-females receiving antiandrogens, GnRH and estrogens which can be associated with serum enzyme elevations but has not been linked to clinically apparent liver injury in transgender women).
Choudhary NS, Bodh V, Chaudhari S, Saraf N, Saigal S. (2017). Norethisterone related drug induced liver injury: a series of 3 cases. J Clin Exp Hepatol. (3 women, ages 27, 43 and 52 with uterine fibroids and vaginal bleeding were treated with norethisterone [5-15 mg daily] for 3-8 weeks when they were found to have abnormal liver tests [bilirubin 0.2-1.0 mg/dL, ALT 614-1058 U/L, Alk P 89-151 U/L], improving within days of stopping the progestin).
Stannov SU, Ries A, Bang UC. (2019). Hepatotoxicity induced by a second-generation combined oral contraceptive: case report and review of the literature. Eur J Contracept Reprod Health Care. (24 year old woman was found to have ALT elevations without jaundice 4 months after starting oral contraceptives [20 mg ethinyl estradiol and 150 µg levonorgestrel] which rose from 156 to 675 U/L until the OCC were stopped, but then arose anew within 2 weeks of restarting [ALT rising from 15 to 109 U/L], again resolving rapidly upon stopping).
Jetter A, Kullak-Ublick GA. (2020). Drugs and hepatic transporters: A review. Pharmacol Res. (Review of the effects of medications on hepatic transporters, mentions that estrogens are substrates for MRP2 which transport them out of the hepatocyte into the canaliculus).

## OTHER REFERENCE LINKS

1 Recent References on Estrogens: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=estrogens/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Estrogens: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=estrogens)